# Sofosbuvir

## OVERVIEW

### Introduction

Sofosbuvir is an oral nucleoside analogue and potent inhibitor of the hepatitis C virus (HCV) RNA polymerase that is used in combination with other antiviral agents to treat chronic hepatitis C. Elevations in serum enzyme levels during sofosbuvir therapy are uncommon, and it has not been implicated convincingly in cases of clinically apparent liver injury with jaundice. Nevertheless, and for unknown reasons, successful antiviral therapy of hepatitis C with sofosbuvir and other direct acting agents in patients with cirrhosis is occasionally complicated by hepatic decompensation; furthermore, treatment can cause reactivation of hepatitis B in susceptible patients coinfected with the hepatitis B virus (HBV).

### Background

Sofosbuvir (soe fos' bue vir) is an orally available nucleotide analogue that has potent activity against the RNA-dependent RNA polymerase of the hepatitis C virus (HCV). Sofosbuvir is a monophosphorylated uracil derivative whose single phosphate is protected by an alaninate cap that allows for the absorption and uptake of the molecule by hepatocytes where it is hydrolyzed to sofosbuvir monophosphate. Intracellular host kinases then convert it to the active triphosphate moiety. In multiple clinical trials, sofosbuvir has been shown to cause a rapid and marked decline in serum HCV RNA levels and, in combination with other antiviral agents and with more prolonged therapy, to result in sustained clearance of HCV (sustained virological response: SVR) in a high proportion of patients. Sofosbuvir was approved for use in the United States in 2013 to be used in combination with ribavirin or with both peginterferon and ribavirin in patients with chronic hepatitis C, genotypes 1, 2, 3 or 4. Sofosbuvir is available in tablets of 400 mg under the brand name Solvaldi, the recommended dose being 400 mg once daily in combination with either ribavirin alone (1000 or 1200 mg daily for 12 weeks for genotype 2 and 24 weeks for genotype 3) or in combination with both ribavirin and peginterferon for 12 weeks for patients with genotype 1.

Subsequently, a fixed combination of sofosbuvir (400 mg) and the HCV NS5A replication complex inhibitor ledipasvir (le dip' as vir: 90 mg) was approved for use in patients with chronic hepatitis C, genotype 1 in 2014 and for genotype 4 in 2015. This combination is available as a fixed dose, single tablet under the brand name Harvoni and the recommended dose is one tablet daily for 12 weeks, which can be shortened to 8 weeks in selected patients.

In addition, sofosbuvir combined with NS5A inhibitors with broader activity against HCV genotypes, daclatasvir (dak lat' as vir: 2015) and velpatasvir (vel pat' as vir: 2016), has been shown to be effective in treating almost all HCV genotypes with sustained response rates of 95% or greater in response to 12 weeks of treatment in genotypes 1, 2, 4, 5 and 6. In 2016, the fixed combination of sofosbuvir (400 mg) and velpatasvir (100 mg) was approved for use in patients with all 6 genotypes of hepatitis C. This combination is available as a fixed dose, single tablet under the brand name Epclusa. The recommended dose is one tablet daily for 12 weeks. For patients with decompensated cirrhosis (Childs-Pugh Class B or C), ribavirin (1000 to 1200 mg in two divided doses daily) should be added to Epclusa for 12 weeks. Finally, the combination of sofosbuvir with an HCV specific NS3/4 protease inhibitor (such as simeprevir [2014]) was also shown to be highly effective in patients with genotype 1 infection generally in 12 week courses.

For patients who fail to respond to a two or three drug combination of direct acting antiviral agents, combinations of potent agents active against the three major HCV polypeptide products have been developed and have shown excellent activity in these refractory patients. The first such regimen was a single tablet formulation of sofosbuvir (400 mg), velpatasvir (100 mg) and a potent, broad spectrum (pangenomic) HCV protease inhibitor, voxilaprevir (100 mg). This combination was approved for use in the United States in 2017 and is available under the brand name Vosevi. The recommended dosing regimen is 1 tablet daily for 12 weeks. This regimen is not recommended for patients with decompensated cirrhosis (Childs-Pugh Class B or C).

As such, sofosbuvir transformed the therapy of chronic hepatitis C and became the most commonly used HCV-specific antiviral agent, replacing peginterferon and combinations of peginterferon, ribavirin and protease inhibitors. Sofosbuvir has few side effects and in placebo controlled trials adverse events occurred at a similar rate with sofosbuvir as placebo. Side effects may include headache, dizziness, nausea and diarrhea. Rare, but potentially severe adverse events include marked bradycardia when sofosbuvir is given with amiodarone.

### Hepatotoxicity

In large randomized controlled trials, serum enzymes elevations were uncommon in patients treated with sofosbuvir despite the fact that the patients being treated had chronic liver disease. In most situations, serum aminotransferase levels improved rapidly upon initiating sofosbuvir therapy, and de novo, late elevations of ALT above 3 times the upper limit of normal (ULN) were uncommon and less frequent than with placebo or no therapy. In multiple, large clinical trials sofosbuvir has not been linked to instances of clinically apparent liver injury with jaundice. Because sofosbuvir is always used with other antiviral agents, it is not always possible to separate the relative role of sofosbuvir from other drugs in causing adverse reactions.

Two rare and unusual forms of liver injury of uncertain relationship to sofosbuvir have been described in patients with receiving antiviral therapy for hepatitis C: sudden hepatic decompensation in patients with preexisting cirrhosis and reactivation of hepatitis B in patients with preexisting evidence of HBV infection.

A rare, but striking liver injury associated with sofosbuvir (and perhaps other potent agents active against HCV) is hepatic decompensation occurring in patients with preexisting cirrhosis. In several instances, decompensation occurred within 2 to 6 weeks of starting therapy (Case 1), while in others it occurred late during therapy or in the immediate posttreatment period. The typical pattern of onset was a progressive rise in bilirubin with signs of hepatic failure such as prolongation of the prothrombin time, decrease in serum albumin and appearance of ascites and hepatic encephalopathy. In many (but not all) instances, serum enzyme levels did not change or increased only slightly in comparison to pretreatment values. In all instances, sofosbuvir was being used in combination with other antiviral agents, such as peginterferon, simeprevir, daclatasvir or ledipasvir, and the specific role of sofosbuvir has been difficult to define. The decompensation usually coincided with rapid viral clearance and patients who survived the episode often had a sustained virological response. The cause of this decompensation is not clear, but it may represent a response to HCV viral eradication (on-target effect) rather than toxicity of the administered antiviral agents (off-target effect on the liver). Alternatively, the injury may be coincidental and unrelated to therapy.

A second form of liver injury that can occur with sofosbuvir therapy and perhaps other potent anti-HCV agents is reactivation of hepatitis B. More than 50 instances of clinically apparent hepatitis with rises in serum HBV DNA levels during therapy of patients for chronic hepatitis C. The majority of these patients were also HBsAg positive with no detectable or only low levels of HBV DNA before treatment (Case 2). Reactivation has also been described in patients who have anti-HBc without HBsAg in serum, a pattern that suggests previous recovery from hepatitis B. HBV reactivation typically arises within 2 to 8 weeks of starting therapy for hepatitis C and it can be clinically manifest with symptoms of acute hepatitis and marked elevations in serum aminotransferase levels and bilirubin. Instances of death from HBV reactivation have been reported with sofosbuvir therapy. The cause of reactivation is unclear, but it may be that HCV replication has a nonspecific suppressive effect on HBV replication, and eradication of HCV allows HBV replication to increase to levels that cause hepatitis. Alternatively, the change in immune reactivity with sudden clearance of HCV or as a result of a direct activity of the antiviral agents may alter the replicative status of HBV.

Likelihood score: A (well known cause of hepatic decompensation in patients with hepatitis C and cirrhosis and a rare cause of reactivation of hepatitis B in susceptible individuals).

### Mechanism of Injury

The mechanism by which sofosbuvir might cause liver injury is not known. It is metabolized in the liver largely via the cytochrome P450 system, predominantly CYP 1A2. Sudden decompensation and the reactivation of HBV during sofosbuvir therapy may reflect changes in the immune status resulting from the suppression of HCV replication and injury.

### Outcome and Management

Therapy of chronic hepatitis C with sofosbuvir is generally well tolerated and has not been linked to serum enzyme elevations or idiosyncratic clinically apparent liver injury. Sofosbuvir in combination with other antiviral agents, however, has been linked to instances of hepatic decompensation in patients with cirrhosis and with rare instances of reactivation of hepatitis B.

In two situations, however, monitoring for liver injury during sofosbuvir therapy is advisable. In patients with advanced cirrhosis, careful monitoring of liver tests during therapy is warranted and treatment discontinued early if progressive rises in serum bilirubin occur in the context of possible hepatic decompensation. Furthermore, patients receiving antiviral therapy for hepatitis C should be screened for evidence of hepatitis B (HBsAg and anti-HBc) before starting therapy. If these virologic markers are present, it is prudent to monitor serum HBV DNA levels, and antiviral therapy for hepatitis B started if viral titers rise. Alternatively, patients may be given prophylaxis against HBV replication for the period of treatment and for 12 weeks of follow up after therapy of hepatitis C. The efficacy of these approaches has not, however, been demonstrated in prospective controlled trials.

Drug Class: Antiviral Agents, Hepatitis C Agents

## CASE REPORTS

### Case 1. Hepatic decompensation during antiviral therapy with sofosbuvir, daclatasvir and ribavirin.(1)

A 74 year old man with chronic hepatitis C, genotype 1a, and advanced cirrhosis and HIV coinfection was started on compassionate use therapy with sofosbuvir (400 mg daily), ledipasvir (90 mg daily) and ribavirin (600 mg twice daily). He was known to have cirrhosis for several years and had a previous episode of decompensation during unsuccessful therapy with peginterferon and ribavirin. He had esophageal varices and ascites which was controlled on spironolactone. His HIV infection was well controlled on efavirenz, tenofovir and emtricitabine which he had taken chronically. Within 2 weeks of starting the oral regimen for hepatitis C, he developed worsening jaundice (Table), and he was admitted for evaluation and therapy for suspected septicemia (piperacillin-tazobactam). He had no rash, fever or eosinophilia. Because of rising bilirubin levels, sofosbuvir, ledipasvir and ribavirin were discontinued. Tests for acute hepatitis A, B and E were negative as were virologic tests for EBV, CMV, HSV and adenovirus infection. Ultrasound and MRCP showed no evidence of biliary obstruction or masses. A liver biopsy showed cirrhosis, marked inflammation and cholestasis which was interpreted as compatible with drug induced liver injury. Lactate levels were normal, but INR levels rose and serum albumin decreased. He continued to worsen, but was not considered a candidate for liver transplantation and died of multiorgan failure and sepsis, 38 days after starting and 20 days after stopping treatment.

#### Key Points

Medication: | Sofosbuvir, ledipasvir, ribavirin
Pattern: | Acute on chronic liver failure
Severity: | Fatal
Latency: | 2 weeks
Recovery: | None
Other medications: | Efavirenz, tenofovir, emtricitabine, spironolactone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 0 | 45 | 204 | 3.7 | INR 1.4, hemoglobin 11.7 g/dL
Day 0 | 0 | 65 | 271 | 5.3 | Therapy started, HCV RNA ~30,000 IU/mL
Day 7 | 0 | 55 | 205 | 7.7 | Hemoglobin 11.4
Day 15 | 0 | 52 | 196 | 16.1 | Admission, hemoglobin 10.1, INR 1.5
Day 18 | 0 | 53 | 202 | 23.5 | Therapy stopped
Day 24 | Day 6 | 50 | 186 | 25.0 | INR 1.9
Day 30 | Day 12 | 50 | 184 | 30.6 | INR 2.4
Day 38 | Day 20 | | | | Died of multiorgan failure
Normal Values | | <40 | <150 | <1.2

#### Comment

An elderly man with partially decompensated cirrhosis due to hepatitis C as well as HIV coinfection developed worsening decompensation when he was started on an all-oral regimen of therapy for hepatitis C. The timing of the clinical worsening was compatible with a drug induced etiology. However, there were several features that did not support the conclusion that therapy was responsible for the decompensation. For one thing, his liver disease seemed to be worsening even before therapy was started, serum bilirubin levels having risen from 3.7 to 5.3 mg/dL. Furthermore, the clinical pattern of injury that arose was unusual in that ALT and Alk P levels did not change, despite the steady increase in serum bilirubin values. Indeed, worsening of the INR did not occur until he was admitted and underwent other therapies and liver biopsy. He also had a history of liver decompensation during previous antiviral therapy with peginterferon and ribavirin, perhaps implicating ribavirin as a cause. While ribavirin regularly causes hemolysis and anemia with rises in serum bilirubin, in this instance hemoglobin levels fell little (from 11.7 to 10.1 g/dL) and the rise in bilirubin was in both direct and indirect fractions. Other evidence of hepatic synthetic dysfunction and liver failure followed. Finally, the patient also had HIV coinfection and was taking 3 other antiviral agents, and the possibility exists of unusual drug-drug interactions. Nevertheless, this and several other cases of hepatic decompensation during successful therapy of HCV related cirrhosis indicate that such patients should be cautioned about this outcome and monitored carefully, particularly during the first month of treatment. The cause of the decompensation is unclear and theoretically may be related to the rapid eradication of HCV infection or change in immune reactivity rather than to a direct hepatotoxic effect of the drug.

### Case 2. Reactivation of hepatitis B during antiviral therapy with sofosbuvir and simeprevir.(2)

A 55 year old man with chronic hepatitis C, genotype 1a, and cirrhosis who also had a history of chronic HBV infection, was started on compassionate use therapy with sofosbuvir (400 mg daily) and simeprevir (dose not given). He was known to have cirrhosis for several years and had previously failed to respond to courses of peginterferon and ribavirin. The cirrhosis was well compensated, but he had evidence of portal hypertension and esophageal varices. Before treatment, HCV RNA levels were 1.3 million IU/mL with serum ALT 62 U/L, bilirubin 0.7 mg/dL, INR 1.05 and platelet count 135,000/μL. Tests for hepatitis B surface antigen (HBsAg) were positive, but hepatitis B e antigen (HBeAg) was negative and antibody to HBeAg (anti-HBe) was present. Serum HBV DNA levels were low but detectable (peak values 2300 IU/mL). Seven weeks into sofosbuvir/simeprevir therapy, the patient developed fatigue, nausea, and abdominal pain followed by dark urine and jaundice. At this point serum ALT was 1495 U/L, AST 1792 U/L, bilirubin 12.2 mg/dL and INR 1.96 (Table). HCV RNA levels, however, were below the level of detection (none). Tests for hepatitis E and HIV infection were negative and autoantibodies were not present. HBV DNA values, however, were high, initially 22 million IU/mL. The drugs for hepatitis C were stopped and he was started on tenofovir and emtricitabine (Truvada). His liver tests began to improve and two months later all tests were normal. HBV DNA levels also fell and became undetectable approximately 4 months after starting treatment for hepatitis B. Fortunately, he remained HCV RNA negative despite having stopped therapy early and was considered to have had a sustained virological response.

#### Key Points

Medication: | Sofosbuvir, simeprevir
Pattern: | Hepatocellular (R ratio not available: no alkaline phosphatase values)
Severity: | Severe (jaundice, hospitalization, rise in INR)
Latency: | 7 weeks
Recovery: | 2 months one
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Bilirubin* (mg/dL) | HCV RNA (IU/mL) | HBV DNA (IU/mL) | Other
Pre | 0 | 62 | 0.7 | | 2300 | INR 1.05
Day 0 | 0 | 60 | 0.9 | 1.3 million | | HCV therapy started
Week 2 | 0 | 30 | 0.5 | 26
Week 4 | 0 | 30 | 0.5 | None
Week 7 | 0 | | | | | Symptomatic
Week 8 | 0 | 1495 | 12.2 | None | | Therapy stopped, INR 1.96
Week 9 | Week 1 | 950 | 19.0 | | 22 million | Tenofovir/emtricitabine
Week 10 | Week 2 | 375 | 13.0 | None
Week 12 | Week 4 | 110 | 3.0 | None | 1000
Week 13 | Week 5 | 70
Week 15 | Week 7 | 30 | 1.5 | None | 100
Week 28 | Week 18 | 30 | 0.5 | None | None
Normal Values | | <40 | <1.2 | None | None

* Some values estimated from Figure 1.

#### Comment

A man with cirrhosis due to hepatitis C who was also a HBsAg carrier with low levels of HBV DNA and no HBeAg in serum was started on oral antiviral therapy for hepatitis C using sofosbuvir and the HCV protease inhibitor simeprevir, a combination that had been shown to be highly effective, although not specifically approved for use at the time. The viral response was prompt, and HCV RNA levels were below the level of detection within 4 weeks of starting treatment. Serum ALT levels also improved. Three weeks later, however, he developed symptoms of hepatitis and was found to have marked, de novo elevations in ALT and bilirubin accompanied by high levels of HBV DNA in serum, indicative of reactivation of chronic hepatitis B. The HCV therapy was stopped and he was started on oral antiviral therapy for hepatitis B (Truvada: the single tablet combination of tenofovir and emtricitabine). He began to improve, and HBV DNA levels gradually fell below his baseline values and were no longer detectable approximately 4 months after starting therapy (decreases in viral levels are much slower in hepatitis B than C). Interestingly, he achieved an SVR, despite stopping HCV therapy early, after only 8 weeks of treatment. Such shortened courses of treatment can be effective, but are not recommended, particularly for patients with cirrhosis. Why treatment of hepatitis C might cause reactivation of an underlying inactive or only minimally active hepatitis B is unknown. However, there is some degree of competition for “replicative space” within hepatocytes between the two viruses–active HCV infection inhibiting HBV replication and vice versa. Thus, reactivation may occur because of loss of the normal inhibitory activity of HCV replication. At least 50 instances of reactivation of hepatitis B during antiviral therapy of hepatitis C have been reported, some of which were fatal. What is unknown is whether reactivation occurs specifically with certain direct acting anti-HCV agents (such as sofosbuvir) or whether it is a general phenomenon that can occur with any potent regimen. Regardless, screening for hepatitis B is recommended before treating patients for hepatitis C, appropriate tests including HBsAg and anti-HBc. Approaches to prevention might be prophylaxis with an anti-HBV agent (tenofovir or entecavir for instance), or early introduction of treatment if HBV DNA levels rise (which requires active monitoring at 4 week intervals). The frequency of reactivation with HCV therapy is unknown but is likely to be uncommon.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sofosbuvir – Sovaldi®

Sofosbuvir/Ledipasvir – Harvoni®

Sofosbuvir/Velpatasvir – Epclusa®

Sofosbuvir/Velpatasvir/Voxilaprevir – Vosevi®

DRUG CLASS

Hepatitis C Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=sofosbuvir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sofosbuvir | 1190307-88-0 | C22-H29-F-N3-O9-P
Ledipasvir | 1256388-51-8 | C49-H54-F2-N8-O6
Velpatasvir | 1377049-84-7 | C49-H54-N8-O8
Voxilaprevir | 1535212-07-7 | C40-H52-F4-N6-O9-S

## CITED REFERENCES

1 Dyson JK, Hutchinson J, Harrison L, Rotimi O, Tiniakos D, Foster GR, Aldersley MA, et al. (2016). Liver toxicity associated with sofosbuvir, an NS5A inhibitor and ribavirin use. J Hepatol.
2 Collins JM, Raphael KL, Terry C, Cartwright EJ, Pillai A, Anania FA, Farley MM., Hepatitis B. (2015). Virus reactivation during successful treatment of hepatitis C virus with sofosbuvir and simeprevir. Clin Infect Dis.

## ANNOTATED BIBLIOGRAPHY

References updated: 07 February 2022

Abbreviations used: HCV, hepatitis C virus; DAA, direct acting antiviral agents; HIV, human immunodeficiency virus; SVR, sustained virological response.

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss oral, direct acting antiviral agents used to treat hepatitis C).
Lohmann V, Körner F, Herian U, Bartenschlager R. (1997). Biochemical properties of hepatitis C virus NS5B RNA-dependent RNA polymerase and identification of amino acid sequence motifs essential for enzymatic activity. J Virol. (Analysis of the biochemical and structural features of the NS5B HCV RNA polymerase and critical regions for its binding to RNA and replicative activity).
Lesburg CA, Cable MB, Ferrari E, Hong Z, Mannarino AF, Weber PC. (1999). Crystal structure of the RNA-dependent RNA polymerase from hepatitis C virus reveals a fully encircled active site. Nat Struct Biol. (Description of the crystal structure of the HCV RNA polymerase [NS5B], which has a unique shape with thumb and fingers subdomains that encircle the template primer and growing RNA chain and allows for design of agents that might inhibit its activity).
Lawitz E, Lalezari JP, Hassanein T, Kowdley KV, Poordad FF, Sheikh AM, Afdhal NH, et al. (2013). Sofosbuvir in combination with peginterferon alfa-2a and ribavirin for non-cirrhotic, treatment-naive patients with genotypes 1, 2, and 3 hepatitis C infection: a randomised, double-blind, phase 2 trial. Lancet Infect Dis. (Among 122 previously untreated patients with chronic hepatitis C, genotypes 1, 2 or 3, who received sofosbuvir [200 or 400 mg daily] or placebo for 12 weeks combined with peginterferon and ribavirin for 12 to 28 weeks, SVR rates were 90-92% with sofosbuvir and 58% with placebo; ALT and AST elevations occurred in 5 patients on sofosbuvir within 4 weeks of starting therapy, remaining elevated during treatment and resolving once peginterferon was stopped).
Kowdley KV, Lawitz E, Crespo I, Hassanein T, Davis MN, DeMicco M, Bernstein DE, et al. (2013). Sofosbuvir with pegylated interferon alfa-2a and ribavirin for treatment-naïve patients with hepatitis C genotype-1 infection (ATOMIC): an open-label, randomised, multicentre phase 2 trial. Lancet. (Among 316 previously treated patients with chronic hepatitis C, genotypes 1, 4, 5 or 6, treated with 12 or 24 weeks with sofosbuvir, peginterferon and ribavirin, SVR rates were 87% to 89%, ALT elevations above 5 times ULN occurred in 4 patients [1%] and 1 patient developed an autoimmune hepatitis, but these abnormalities were attributed to peginterferon).
Jacobson IM, Gordon SC, Kowdley KV, Yoshida EM, Rodriguez-Torres M, Sulkowski MS, Shiffman ML, et al. (2013). POSITRON Study; FUSION Study. Sofosbuvir for hepatitis C genotype 2 or 3 in patients without treatment options. N Engl J Med. (Among 278 patients with chronic hepatitis C, genotypes 2 and 3, treated in two trials of sofosbuvir and ribavirin for 12 or 16 weeks or placebo for 12 weeks, the overall SVR rate was 78% vs 0% with placebo; serious adverse events occurred in 3% of placebo and 3% to 5% of sofosbuvir-ribavirin recipients, only one patient(on placebo) discontinuing therapy early for liver related issues: ALT elevations).
Lawitz E, Mangia A, Wyles D, Rodriguez-Torres M, Hassanein T, Gordon SC, Schultz M, et al. (2013). Sofosbuvir for previously untreated chronic hepatitis C infection. N Engl J Med. (Two trials of sofosbuvir in patients with chronic hepatitis C; among 327 with genotype 1,4,5 or 6 infection treated with 12 weeks of sofosbuvir, peginterferon and ribavirin, the SVR rate was 90%; among 499 with genotype 2 or 3 infection treated with sofosbuvir and ribavirin for 12 vs peginterferon and ribavirin for 24 weeks, the SVR rate was 67% in both groups; adverse events were more frequent in peginterferon treated groups and no patient on sofosbuvir required discontinuation because of ALT elevations or liver related adverse events).
Osinusi A, Meissner EG, Lee YJ, Bon D, Heytens L, Nelson A, Sneller M, et al. (2013). Sofosbuvir and ribavirin for hepatitis C genotype 1 in patients with unfavorable treatment characteristics: a randomized clinical trial. JAMA. (Among 60 previously untreated patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and ribavirin [1000-1200 or 600 mg daily], SVR rates were 68% with standard ribavirin doses [1000-1200 mg daily] and 47% with low doses [600 mg daily]; there were no serious adverse events requiring drug discontinuation).
Lawitz E, Poordad FF, Pang PS, Hyland RH, Ding X, Mo H, Symonds WT, et al. (2014). Sofosbuvir and ledipasvir fixed-dose combination with and without ribavirin in treatment-naive and previously treated patients with genotype 1 hepatitis C virus infection (LONESTAR): an open-label, randomised, phase 2 trial. Lancet. (Among 100 patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir with or without ribavirin for 8 or 12 weeks, SVR rates were 95% to 100%, all serious adverse events related to therapy were attributed to ribavirin and there were no de novo ALT elevations).
Sulkowski MS, Gardiner DF, Rodriguez-Torres M, Reddy KR, Hassanein T, Jacobson I, Lawitz E, et al. (2014). AI444040 Study Group. Daclatasvir plus sofosbuvir for previously treated or untreated chronic HCV infection. N Engl J Med. (Among 211 patients with chronic hepatitis C treated with sofosbuvir and daclatasvir with or without ribavirin for 24 weeks, SVR rates were 98% [genotype 1], 92% [genotype 2] and 89% [genotype 3]; most adverse events were fatigue, headache and nausea, and there were no ALT elevations above 5 times ULN or liver related serious adverse events).
Pellicelli AM, Montalbano M, Lionetti R, Durand C, Ferenci P, D'Offizi G, Knop V, et al. (2014). Sofosbuvir plus daclatasvir for post-transplant recurrent hepatitis C: potent antiviral activity but no clinical benefit if treatment is given late. Dig Liver Dis. (Among 12 patients with severe chronic hepatitis C, genotype 1 and 4, after liver transplantation treated with sofosbuvir and daclatasvir with or without ribavirin for 24 weeks, 3 died of progressive hepatic failure during therapy [weeks 4, 8 and 10] and the other 9 had an SVR).
Gane EJ, Stedman CA, Hyland RH, Ding X, Svarovskaia E, Subramanian GM, Symonds WT, et al. (2014). Efficacy of nucleotide polymerase inhibitor sofosbuvir plus the NS5A inhibitor ledipasvir or the NS5B non-nucleoside inhibitor GS-9669 against HCV genotype 1 infection. Gastroenterology. (Among 113 patients with chronic hepatitis C, genotype 1, treated with various combinations of sofosbuvir, ledipasvir, ribavirin and an NS5B non-nucleoside inhibitor for 6-12 weeks, SVR rates were excellent with all regimens, and there were no liver related adverse events).
Afdhal N, Zeuzem S, Kwo P, Chojkier M, Gitlin N, Puoti M, Romero-Gomez M, et al. (2014). ION-1 Investigators. Ledipasvir and sofosbuvir for untreated HCV genotype 1 infection. N Engl J Med. (Among 865 patients with previously untreated chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir [with or without ribavirin] for 12 or 24 weeks, SVR rates were high in all groups [97% to 99%] and side effects were generally mild; no patient developed a liver related serious adverse event; no mention of ALT elevations).
Afdhal N, Reddy KR, Nelson DR, Lawitz E, Gordon SC, Schiff E, Nahass R, et al. (2014). ION-2 Investigators. Ledipasvir and sofosbuvir for previously treated HCV genotype 1 infection. N Engl J Med. (Among 440 patients with previously treated chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir with or without ribavirin, SVR rates were higher with 24 weeks [99% and 99%] than 12 weeks [94% and 96%] of combination therapy regardless of addition of ribavirin, and adverse events were generally mild without ribavirin therapy, no patient requiring early discontinuation, although one patient developed hepatic encephalopathy).
Kowdley KV, Gordon SC, Reddy KR, Rossaro L, Bernstein DE, Lawitz E, Shiffman ML, et al. (2014). ION-3 Investigators. Ledipasvir and sofosbuvir for 8 or 12 weeks for chronic HCV without cirrhosis. N Engl J Med. (Among 647 previously untreated, noncirrhotic patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir [with or without ribavirin] for 8 or 12 weeks, SVR rates were high in all groups [93% to 95%]; ALT elevations occurred in 5 patients [<1%] and were above 5 times ULN in 1, but no patient required early discontinuation for a liver related adverse event).
Hoofnagle JH, Sherker AH. (2014). Therapy for hepatitis C--the costs of success. N Engl J Med. (Editorial in response to results of three controlled trials of sofosbuvir and ledipasvir in chronic hepatitis C [Afdhal 2014, Afdhal 2014, Kowdley 2014]).
Zeuzem S, Dusheiko GM, Salupere R, Mangia A, Flisiak R, Hyland RH, Illeperuma A, et al. (2014). VALENCE Investigators. Sofosbuvir and ribavirin in HCV genotypes 2 and 3. N Engl J Med. (Among 419 patients with chronic hepatitis C treated with varying regimens of sofosbuvir with ribavirin or placebo for 12 weeks [genotype 2] or sofosbuvir with ribavirin for 12 or 24 weeks [genotype 3], highest SVR rates were achieved with 12 weeks in genotype 2 [93%] and 24 weeks in genotype 3 patients [85%]; no serious liver related adverse events were reported among patients receiving therapy).
Lawitz E, Sulkowski MS, Ghalib R, Rodriguez-Torres M, Younossi ZM, Corregidor A, DeJesus E, et al. (2014). Simeprevir plus sofosbuvir, with or without ribavirin, to treat chronic infection with hepatitis C virus genotype 1 in non-responders to pegylated interferon and ribavirin and treatment-naïve patients: the COSMOS randomised study. Lancet. (Among 167 patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir [with or without ribavirin] for 12 or 24 weeks, SVR rates were 90% to 94%; no mention of ALT elevations or hepatotoxicity).
Sulkowski MS, Naggie S, Lalezari J, Fessel WJ, Mounzer K, Shuhart M, Luetkemeyer AF, et al. (2014). PHOTON-1 Investigators. Sofosbuvir and ribavirin for hepatitis C in patients with HIV coinfection. JAMA. (Among 223 patients with chronic hepatitis C and HIV coinfection treated with sofosbuvir and ribavirin for 12 or 24 weeks, SVR rates ranged from 75-92%; hyperbilirubinemia attributed to ribavirin was most marked in patients also receiving atazanavir for HIV infection).
Omata M, Nishiguchi S, Ueno Y, Mochizuki H, Izumi N, Ikeda F, Toyoda H, et al. (2014). Sofosbuvir plus ribavirin in Japanese patients with chronic genotype 2 HCV infection: an open-label, phase 3 trial. J Viral Hepat. (Among 153 Japanese patients with chronic hepatitis C, genotype 2, treated with sofosbuvir and ribavirin for 12 weeks, the SVR rate was 97% and there were no serious adverse events attributed to sofosbuvir; no mention of ALT elevations or hepatotoxicity).
(2014). A combination of ledipasvir and sofosbuvir (Harvoni) for hepatitis C. Med Lett Drugs Ther. (Concise summary of the pharmacology, clinical efficacy, safety and costs of the fixed combination of ledipasvir and sofosbuvir in chronic hepatitis C, genotype 1; adverse events include headache, fatigue, nausea, diarrhea and insomnia, but there was no comparison to placebo therapy and the relationship of these nonspecific symptoms to the drugs is unclear).
Charlton M, Gane E, Manns MP, Brown RS, Curry MP, Kwo PY, Fontana RJ, et al. (2015). Sofosbuvir and ribavirin for treatment of compensated recurrent hepatitis C virus infection after liver transplantation. Gastroenterology. (Among 40 patients with recurrent, compensated chronic hepatitis C after liver transplantation, who were treated with sofosbuvir and ribavirin for 24 weeks, 70% achieved an SVR and 30% relapsed; but there were no serious adverse events attributed to sofosbuvir and no case of hepatic decompensation).
Lawitz E, Poordad F, Brainard DM, Hyland RH, An D, Dvory-Sobol H, Symonds WT, et al. (2015). Sofosbuvir with peginterferon-ribavirin for 12 weeks in previously treated patients with hepatitis C genotype 2 or 3 and cirrhosis. Hepatology. (Among 47 previously treated patients with chronic hepatitis C, genotype 2 or 3, treated with 12 weeks of sofosbuvir, peginterferon and ribavirin, SVR rates were 89%; one patient developed hepatic decompensation which was attributed to peginterferon).
Pearlman BL, Ehleben C, Perrys M. (2015). The combination of simeprevir and sofosbuvir is more effective than that of peginterferon, ribavirin, and sofosbuvir for patients with hepatitis C-related Child's class A cirrhosis. Gastroenterology. (Among 82 patients with chronic hepatitis C and compensated cirrhosis, genotype 1a, who were treated with sofosbuvir and either simeprevir or peginterferon with ribavirin for 12 weeks, SVR rates were higher with simeprevir [93% vs 75%]; one patient on sofosbuvir with peginterferon developed hepatic decompensation, but there were no other liver related serious adverse events).
Nelson DR, Cooper JN, Lalezari JP, Lawitz E, Pockros PJ, Gitlin N, Freilich BF, et al., ALLY-3 Study Team. (2015). All-oral 12-week treatment with daclatasvir plus sofosbuvir in patients with hepatitis C virus genotype 3 infection: ALLY-3 phase III study. Hepatology. (Among 152 patients with chronic hepatitis C, genotype 3, treated with sofosbuvir and daclatasvir for 12 weeks, 135 [89%] had an SVR, and there were no treatment related serious adverse events, early discontinuations for adverse events or de novo ALT elevations above 5 times ULN).
Rodriguez-Torres M, Gaggar A, Shen G, Kirby B, Svarovskaia E, Brainard D, Symonds WT, et al. (2015). Sofosbuvir for chronic hepatitis C virus infection genotype 1-4 in patients coinfected with HIV. J Acquir Immune Defic Syndr. (Among 61 patients with chronic hepatitis C and HIV coinfection who underwent studies of drug interactions with sofosbuvir, no significant changes in pharmacokinetics of antiretroviral agents were found).
Molina JM, Orkin C, Iser DM, Zamora FX, Nelson M, Stephan C, Massetto B, et al. (2015). PHOTON-2 study team. Sofosbuvir plus ribavirin for treatment of hepatitis C virus in patients co-infected with HIV (PHOTON-2): a multicentre, open-label, non-randomised, phase 3 study. Lancet. (Among 274 patients with chronic hepatitis C [genotype 1 to 4] and HIV coinfection treated with sofosbuvir and ribavirin for 12 or 24 weeks, SVR rates were 84% to 89%, common adverse events were fatigue, insomnia, asthenia and headache, serious adverse events occurred in 15 [5%], 4 considered related to therapy, but not to sofosbuvir).
Pungpapong S, Aqel B, Leise M, Werner KT, Murphy JL, Henry TM, Ryland K, et al. (2015). Multicenter experience using simeprevir and sofosbuvir with or without ribavirin to treat hepatitis C genotype 1 after liver transplant. Hepatology. (Among 123 patients with recurrent chronic hepatitis C, genotype 1, after liver transplant who were treated with simeprevir and sofosbuvir with or without ribavirin for 12 weeks, the overall SVR rate was 90% and severe side effects included acute pancreatitis, allergic lung injury and acute urinary obstruction; there were no ALT elevations above 5 times ULN or clinically apparent liver injury).
Cornella SL, Stine JG, Kelly V, Caldwell SH, Shah NL. (2015). Persistence of mixed cryoglobulinemia despite cure of hepatitis C with new oral antiviral therapy including direct-acting antiviral sofosbuvir: A case series. Postgrad Med. (Among 5 patients with chronic hepatitis C and cryoglobulinemia, successful therapy with antiviral regimens resulted in loss of cryoglobulins in only 2 patients and most had persistence of renal and neurologic symptoms despite clearance of virus and resolution of liver disease).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but all were antiretroviral agents and no case was attributed to the oral direct acting agents used to treat hepatitis C).
Bourlière M, Bronowicki JP, de Ledinghen V, Hézode C, Zoulim F, Mathurin P, Tran A, et al. (2015). Ledipasvir-sofosbuvir with or without ribavirin to treat patients with HCV genotype 1 infection and cirrhosis non-responsive to previous protease-inhibitor therapy: a randomised, double-blind, phase 2 trial (SIRIUS). Lancet Infect Dis. (Among 155 previously treated, cirrhotic patients with chronic hepatitis C treated with placebos for 12 weeks followed by sofosbuvir and ledipasvir and ribavirin for 12 weeks vs sofosbuvir and ledipasvir alone for 24 weeks, SVR rates were 96% and 97%; adverse events more frequent on antiviral therapy than occurred during the 12 weeks of placebo therapy included headache, fatigue, irritability, diarrhea and cough, but significant ALT elevations occurred more frequently on placebo [n=7, 9%] than active therapy [n=1, 0.7%]).
Reddy KR, Bourlière M, Sulkowski M, Omata M, Zeuzem S, Feld JJ, Lawitz E, et al. (2015). Ledipasvir and sofosbuvir in patients with genotype 1 hepatitis C virus infection and compensated cirrhosis: An integrated safety and efficacy analysis. Hepatology. (Among 513 cirrhotic patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir with or without ribavirin for 12 or 24 weeks in 7 clinical trials, the overall SVR rate was 96% and there were 24 [5%] serious adverse events, only 5 [1%] of which were considered treatment related, none of which were liver related).
Wyles D, Pockros P, Morelli G, Younes Z, Svarovskaia E, Yang JC, Pang PS, et al. (2015). Ledipasvir-sofosbuvir plus ribavirin for patients with genotype 1 hepatitis C virus previously treated in clinical trials of sofosbuvir regimens. Hepatology. (Among 51 patients with chronic hepatitis C who had failed to respond to a sofosbuvir based regimen and were then treated with sofosbuvir, ledipasvir and ribavirin for 12 weeks, the SVR rate was 98% and there were no severe elevations in serum ALT levels or liver related serious adverse events).
Gutierrez JA, Carrion AF, Avalos D, O'Brien C, Martin P, Bhamidimarri KR, Peyton A. (2015). Sofosbuvir and simeprevir for treatment of hepatitis C virus infection in liver transplant recipients. Liver Transpl. (Among 61 patients with recurrent hepatitis C after liver transplantation who were treated with simeprevir and sofosbuvir for 12 weeks, the overall SVR rate was 93%, two patients with cirrhosis developed hepatic decompensation, but no patient died or had hepatic rejection).
(2015). In brief: severe bradycardia with sofosbuvir and amiodarone. Med Lett Drugs Ther. (Summary of FDA warning regarding life threatening bradycardia in patients on amiodarone therapy who are treated with sofosbuvir, occurring within hours to up to 12 days after starting; 3 patients required pacemakers and one died).
Mizokami M, Yokosuka O, Takehara T, Sakamoto N, Korenaga M, Mochizuki H, Nakane K, et al. (2015). Ledipasvir and sofosbuvir fixed-dose combination with and without ribavirin for 12 weeks in treatment-naive and previously treated Japanese patients with genotype 1 hepatitis C: an open-label, randomised, phase 3 trial. Lancet Infect Dis. (Among 341 Japanese patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir with or without ribavirin for 12 weeks, SVR rates were 98% and 100%, adverse events were more common in those receiving ribavirin [75% vs 65%]; there were no liver related severe adverse events attributed to therapy or ALT elevations above 5 times ULN).
Alqahtani SA, Afdhal N, Zeuzem S, Gordon SC, Mangia A, Kwo P, Fried M, et al. (2015). Safety and tolerability of ledipasvir/sofosbuvir with and without ribavirin in patients with chronic hepatitis C virus genotype 1 infection: Analysis of phase III ION trials. Hepatology. (Among 1952 patients with chronic hepatitis C, genotype 1, enrolled in 3 clinical trials and treated with sofosbuvir and ledipasvir with [n=872] or without [n=1080] ribavirin, adverse events were more frequent in those receiving ribavirin [71% vs 45%] and severe adverse events requiring discontinuation were similar in frequency [0.7% vs 1%]; no mention of ALT elevations or hepatic decompensation).
Charlton M, Everson GT, Flamm SL, Kumar P, Landis C, Brown RS, Fried MW, et al. (2015). SOLAR-1 Investigators. Ledipasvir and sofosbuvir plus ribavirin for treatment of HCV infection in patients with advanced liver disease. Gastroenterology. (Among 337 patients with chronic hepatitis C, genotype 1 or 4, with decompensated cirrhosis treated with sofosbuvir, ledipasvir and ribavirin for 12 or 24 weeks, SVR rates were 86% to 89%, but serious adverse events were frequent [23%] and included hepatic decompensation, need for liver transplantation and death [2.6%]).
Saxena V, Nyberg L, Pauly M, Dasgupta A, Nyberg A, Piasecki B, Winston B, et al. (2015). Safety and Efficacy of simeprevir/sofosbuvir in hepatitis C-infected patients with compensated and decompensated cirrhosis. Hepatology. (Among 156 patients with chronic hepatitis C, genotype 1, and cirrhosis treated with simeprevir and sofosbuvir with or without ribavirin for 12 weeks, overall SVR rates were 91% in compensated vs 73% in decompensated cases, and worsening decompensation in 20% vs 3%, one patient dying of liver failure, but rates of adverse events were said to be similar to those of a matched cohort of untreated subjects).
Leroy V, Dumortier J, Coilly A, Sebagh M, Fougerou-Leurent C, Radenne S, Botta D, et al. (2015). Agence Nationale de Recherches sur le SIDA et les Hépatites Virales CO23 Compassionate Use of Protease Inhibitors in Viral C in Liver Transplantation Study Group. Efficacy of sofosbuvir and daclatasvir in patients with fibrosing cholestatic hepatitis C after liver transplantation. Clin Gastroenterol Hepatol. (Among 23 patients with fibrosing cholestatic hepatitis C after liver transplant treated with sofosbuvir and daclatasvir [n=15] or sofosbuvir and ribavirin [n=8] for 24 weeks, SVR was achieved in 22 [96%]; one patient developed worsening cholestasis after 12 weeks that did not improve when daclatsavir was stopped [16 weeks], but did when sofosbuvir was stopped [24 weeks]).
Fazel Y, Lam B, Golabi P, Younossi Z. (2015). Safety analysis of sofosbuvir and ledipasvir for treating hepatitis C. Expert Opin Drug Saf. (Review of the adverse events and safety of sofosbuvir and ledipasvir in treating chronic hepatitis C including patients with cirrhosis and clinical decompensation).
Collins JM, Raphael KL, Terry C, Cartwright EJ, Pillai A, Anania FA, Farley MM. (2015). Hepatitis B virus reactivation during successful treatment of hepatitis C virus with sofosbuvir and simeprevir. Clin Infect Dis. (2 cases: 55 year old man with chronic hepatitis C, genotype 1, and HBsAg with low levels of HBV DNA [2300 IU/mL] developed jaundice 8 weeks after starting sofosbuvir and simeprevir [bilirubin 12.2 mg/dL, ALT 1495 U/L, INR 1.96, HBV DNA 22 million IU/mL], with resolution within 6 weeks of stopping HCV agents and starting tenofovir and emtricitabine; [Case 2], 57 year old man with chronic hepatitis C, genotype 1a, and anti-HBc without HBsAg developed rising levels of HBV DNA during therapy with sofosbuvir and simeprevir [Pre <20, 2 weeks 353 and 4 weeks 11,255 IU/mL], which fell to undetectable levels within 8 weeks of starting tenofovir with emtricitabine [Truvada], ALT values remaining normal during the episode).
Aqel BA, Pungpapong S, Leise M, Werner KT, Chervenak AE, Watt KD, Murphy JL, et al. (2015). Multicenter experience using simeprevir and sofosbuvir with or without ribavirin to treat hepatitis C genotype 1 in patients with cirrhosis. Hepatology. (Among 119 cirrhotic patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir with or without ribavirin for 12 weeks, SVR was achieved in 78%; bilirubin levels rose above 3 mg/dL in 4 patients, but no patient developed hepatic decompensation on therapy or had to discontinue treatment early because of liver related adverse events; one patient died of liver failure 6 weeks after completing treatment despite having cleared HCV RNA).
Ferenci P, Kozbial K, Mandorfer M, Hofer H. (2015). HCV targeting of patients with cirrhosis. J Hepatol. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis, suggests that genotype 1 infected patients should receive an all-oral regimen such as dual therapy with sofosbuvir and ledipasvir or daclatasvir or the triple combination of dasabuvir with ombitasvir and paritaprevir, the major unresolved issues being duration of therapy and the role of ribavirin).
Backus LI, Belperio PS, Shahoumian TA, Loomis TP, Mole LA. (2015). Effectiveness of sofosbuvir-based regimens in genotype 1 and 2 hepatitis C virus infection in 4026 U.S. Veterans. Aliment Pharmacol Ther. (Analysis outcomes of treatment of 4026 patients with chronic hepatitis C using sofosbuvir based regimens in the Veterans Administration hospitals found relatively low SVR rates, interpreted as representing “real-world” experience rather than selection and management of patients; no mention of adverse events).
Kalafateli M, Dusheiko G, Manousou P. (2015). Clinical decompensation after achieving SVR with sofosbuvir, daclatasvir and ribavirin in a patient with recurrent HCV post-liver transplant. J Gastrointestin Liver Dis. (33 year old man with hemophilia and chronic hepatitis C, genotype 3, underwent liver transplantation and had recurrence of hepatitis C which failed to respond to several courses of peginterferon, eventually achieving an SVR with sofosbuvir, daclatasvir and ribavirin, but then developing hepatic decompensation 2 months later).
Bailly F, Pradat P, Virlogeux V, Zoulim F. (2015). Antiviral therapy in patients with hepatitis C virus-induced cirrhosis. Dig Dis. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis summarizing the high rate of adverse events including hepatic decompensation and death with peginterferon based regimens combined with boceprevir or telaprevir and the more effective and better tolerated all oral regimens).
Kohli A, Kapoor R, Sims Z, Nelson A, Sidharthan S, Lam B, Silk R, et al. (2015). Ledipasvir and sofosbuvir for hepatitis C genotype 4: a proof-of-concept, single-centre, open-label phase 2a cohort study. Lancet Infect Dis. (Among 21 patients with chronic hepatitis C, genotype 4, treated with ledipasvir and sofosbuvir for 12 weeks, 20 [95%] had an SVR and there were no serious adverse events and no mention was made of significant ALT elevations).
Wyles DL, Ruane PJ, Sulkowski MS, Dieterich D, Luetkemeyer A, Morgan TR, Sherman KE, et al. (2015). ALLY-2 Investigators. Daclatasvir plus sofosbuvir for HCV in patients coinfected with HIV-1. N Engl J Med. (Among 203 patients with chronic hepatitis C, genotype 1 to 4, and HIV coinfection treated with sofosbuvir and daclatasvir for 8 or 12 weeks, SVR rates were 97 to 98% [12 weeks] and 76% [8 weeks], and there were no discontinuations for adverse events, treatment related serious adverse events or ALT elevations above 3 times ULN).
Naggie S, Cooper C, Saag M, Workowski K, Ruane P, Towner WJ, Marks K, et al. (2015). ION-4 Investigators. Ledipasvir and sofosbuvir for HCV in patients coinfected with HIV-1. N Engl J Med. (Among 335 patients with chronic hepatitis C, genotype 1 or 4, and HIV coinfection who were treated with sofosbuvir and ledipasvir for 12 weeks while maintained on antiretroviral therapy, 322 [96%] had an SVR and serious adverse events occurred in 8 patients [2%] which included 2 cases of hepatocellular carcinoma, 2 portal vein thrombosis and 3 serious infections, one of which was fatal [endocarditis]; ALT elevations above 5 times ULN occurred in only 1 patient [0.3%]).
Renet S, Chaumais MC, Antonini T, Zhao A, Thomas L, Savoure A, Samuel D, et al. (2015). Extreme bradycardia after first doses of sofosbuvir and daclatasvir in patients receiving amiodarone: 2 cases including a rechallenge. Gastroenterology. (Two patients taking amiodarone developed severe bradycardia within 2 hours of receiving sofosbuvir and daclatasvir, one with recurrence upon restarting therapy 13 days, but not 8 weeks after stopping the amiodarone).
Shiffman ML, James AM, Long AG, Alexander PC. (2015). Treatment of chronic HCV with sofosbuvir and simeprevir in patients with cirrhosis and contraindications to interferon and/or ribavirin. Am J Gastroenterol. (Among 120 cirrhotic patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir for 12 weeks, the SVR rate was 83%, but 14 patients developed complications of cirrhosis including hyperbilirubinemia in 8, sepsis in 2 [1 dying of multiorgan failure], hepatocellular carcinoma in 2 and variceal hemorrhage in 2).
Ende AR, Kim NH, Yeh MM, Harper J, Landis CS. (2015). Fulminant hepatitis B reactivation leading to liver transplantation in a patient with chronic hepatitis C treated with simeprevir and sofosbuvir: a case report. J Med Case Rep. (59 year old woman with chronic hepatitis C, genotype 1, and anti-HBc without HBsAg or HBV DNA in serum, developed jaundice 11 weeks after starting sofosbuvir and simeprevir [bilirubin 9.1 mg/dL, ALT 2263 U/L, INR 1.9, HBV DNA 29 million IU/mL]; she was started on tenofovir, but developed progressive liver failure and underwent emergency liver transplantation 10 days after presentation).
Lawitz E, Jacobson IM, Nelson DR, Zeuzem S, Sulkowski MS, Esteban R, Brainard D, et al. (2015). Development of sofosbuvir for the treatment of hepatitis C virus infection. Ann N Y Acad Sci. (Review of the development of therapy of hepatitis C, focusing upon sofosbuvir and the prelicensure studies that lead to its approval).
Gane EJ, Hyland RH, An D, Svarovskaia E, Pang PS, Brainard D, Stedman CA. (2015). Efficacy of ledipasvir and sofosbuvir, with or without ribavirin, for 12 weeks in patients With HCV genotype 3 or 6 infection. Gastroenterology. (Among 101 patients with chronic hepatitis C genotype 3 and 25 with genotype 6 who were treated with sofosbuvir and ledipasvir with or without ribavirin for 12 weeks, SVR rates were 64% to 100% with genotype 3 and 96% with genotype 6; serious adverse events occurred in 6 patients [5%], but only 1 led to stopping therapy, none were liver related and no patient died).
Foster GR, Pianko S, Brown A, Forton D, Nahass RG, George J, Barnes E, et al., BOSON Study Group. (2015). Efficacy of sofosbuvir plus ribavirin with or without peginterferon-alfa in patients with hepatitis C virus genotype 3 infection and treatment-experienced patients with cirrhosis and hepatitis C virus genotype 2 infection. Gastroenterology. (Among 592 patients with chronic hepatitis C, genotype 2 or 3, treated with sofosbuvir and ribavirin for 16 or 24 weeks or sofosbuvir, ribavirin and peginterferon for 12 weeks, the SVR rates were 87% to 100% in genotype 2 and 71% to 93% in genotype 3 patients; serious adverse events occurred in 4% to 6%, but none were hepatic decompensation or hepatitis and most were considered unrelated to sofosbuvir; ALT elevations above 5 times ULN occurred in 9 patients [1.5%], but were self-limited and did not result in early discontinuation of therapy).
European Association for Study of Liver. (2015). EASL Recommendations on Treatment of Hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver disease research and academic society).
AASLD/IDSA HCV Guidance Panel. (2015). Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies).
Feld JJ, Jacobson IM, Hezode C, Asselah T, Ruane PJ, Gruener N, Abergel A, et al. (2015). Sofosbuvir and velpatasvir for HCV genotype 1, 2, 4, 5 and 6 infection. N Engl J Med. (Among 741 patients with chronic hepatitis C, genotype 1, 2, 4, 5, or 6, who were treated with a placebo [n=91] vs a single tablet, fixed combination of sofosbuvir and velpatasvir [n=624] once daily for 12 weeks, SVR rates were 0% vs 99% and serious adverse events occurred in none vs 2% on antiviral therapy, but no patient had a liver related serious adverse event or death).
Foster GR, Afdhal N, Roberts SK, Brau N, Gane EJ, Pianko S, Lawitz E, et al. (2015). Sofosbuvir and velpatasvir for HCV genotype 2 and 3 infection. N Engl J Med. (Among 266 patients with chronic hepatitis C, genotype 2 treated with sofosbuvir and velpatasvir vs ribavirin for 12 weeks, SVR rates were 99% vs 94% and adverse events were similar; among 544 patients with genotype 3 infection treated with sofosbuvir and velpatasvir for 12 weeks vs sofosbuvir and ribavirin for 24 weeks, the SVR rates were 97% vs 82%; adverse events were more frequent with ribavirin and no patient had a liver related serious adverse event or death).
Curry MP, O’Leary JG, Bzowej N, Muir AJ, Korenblat KM, Fenkel JM, Reddy R, Lawitz E, et al. (2015). Sofosbuvir and velpatasvir for HCV in patients with decompensated cirrhosis. N Engl J Med. (Among 267 patients with chronic hepatitis C and decompensated cirrhosis who were treated with sofosbuvir and velpatasvir for 12 or 24 weeks vs the combination with ribavirin for 12 weeks, SVR rates ranged from 83% to 94%; serious adverse events occurred in 18%, early discontinuation in 3% and death in 3% [4 from sepsis and 2 liver failure]).
Stedman CA, Hyland RH, Ding X, Pang PS, McHutchison JG, Gane EJ. (2016). Once daily ledipasvir/sofosbuvir fixed-dose combination with ribavirin in patients with inherited bleeding disorders and hepatitis C genotype 1 infection. Haemophilia. (Among 14 patients with an inherited bleeding disorder and chronic hepatitis C, genotype 1, treated with sofosbuvir, lepidasvir and ribavirin for 12 weeks, all had an SVR and none developed a serious liver related or hematologic adverse event).
Everson GT, Towner WJ, Davis MN, Wyles DL, Nahass RG, Thuluvath PJ, Etzkorn K, et al. (2015). Sofosbuvir With Velpatasvir in Treatment-Naive Noncirrhotic Patients With Genotype 1 to 6 Hepatitis C Virus Infection: A Randomized Trial. Ann Intern Med. (Among 377 patients with chronic hepatitis C, genotype 1 or 6, treated with sofosbuvir and velpatasvir [25 or 200 mg] for 12 weeks with or without ribavirin, 337 [89%] had an SVR, and there were no serious liver related adverse events).
Lawitz E, Matusow G, DeJesus E, Yoshida EM, Felizarta F, Ghalib R, Godofsky E, et al. (2016). Simeprevir plus sofosbuvir in patients with chronic hepatitis C virus genotype 1 infection and cirrhosis: A Phase 3 study (OPTIMIST-2). Hepatology. (Among 103 patients with chronic hepatitis C, genotype 1, and cirrhosis treated with sofosbuvir and simeprevir for 12 weeks 103 [83%] had an SVR, and no patient developed liver failure or a treatment related serious adverse event).
Kamar N, Marion O, Rostaing L, Cointault O, Ribes D, Lavayssière L, Esposito L, et al. (2016). Efficacy and safety of sofosbuvir-based antiviral therapy to treat hepatitis C virus infection after kidney transplantation. Am J Transplant. (Among 25 kidney transplant recipients with chronic hepatitis C, genotype 1, treated with sofosbuvir in combination with other antiviral agents, 22 [88%] had an SVR, and "no adverse event was observed").
Sulkowski MS, Vargas HE, Di Bisceglie AM, Kuo PA, Reddy KR, Lim JK, Morelli G, et al., HCV-TARGET Study Group. (2016). Effectiveness of simeprevir plus sofosbuvir, with or without ribavirin, in real-world patients with HCV genotype 1 infection. Gastroenterology. (Among 836 patients with chronic hepatitis C, genotype 1, enrolled in a observational cohort study and treated with sofosbuvir and simeprevir [169 with ribavirin] for up to 16 weeks, the SVR rate was 84% and serious adverse events occurred in 44 patients [5%], with hepatic decompensation in 10 [1.2%], serious infections in 9 [1.1%] and death in 5 [0.6%], 2 attributed to hepatic failure).
Lai CL, Wong VW, Yuen MF, Yang JC, Knox SJ, Mo H, Han LL, et al. (2016). Sofosbuvir plus ribavirin for the treatment of patients with chronic genotype 1 or 6 hepatitis C virus infection in Hong Kong. Aliment Pharmacol Ther. (Among 31 Chinese patients with chronic hepatitis C, genotype 1 or 6, treated with sofosbuvir and ribavirin for 12, 16 or 24 weeks, 30 [97%] had an SVR and none had a serious adverse events or stopped therapy early for therapy related side effects).
Zeng QL, Li CX, Zhang DW, Li W, Xu GH, Yu ZJ. (2016). Letter: safety and efficacy of sofosbuvir plus daclatasvir with ribavirin for 12 weeks in Chinese treatment-experienced cirrhotic genotype 1b patients with HCV. Aliment Pharmacol Ther. (Among 31 patients with chronic hepatitis C and cirrhosis treated with sofosbuvir and daclatasvir for 12 weeks, 30 [97%] had an SVR, and no patient had a serious adverse event or stopped therapy early).
Crittenden NE, Buchanan LA, Pinkston CM, Cave B, Barve A, Marsano L, McClain CJ, et al. (2016). Simeprevir and sofosbuvir with or without ribavirin to treat recurrent genotype 1 hepatitis C virus infection after orthotopic liver transplantation. Liver Transpl. (Among 56 patients with recurrent hepatitis C after liver transplantation who were treated with sofosbuvir and simeprevir for 12 weeks, 49 [88%] had an SVR, and two died of liver failure).
Manns M, Samuel D, Gane EJ, Mutimer D, McCaughan G, Buti M, Prieto M, et al., SOLAR-2 investigators. (2016). Ledipasvir and sofosbuvir plus ribavirin in patients with genotype 1 or 4 hepatitis C virus infection and advanced liver disease: a multicentre, open-label, randomised, phase 2 trial. Lancet Infect Dis. (Among 296 patients with chronic hepatitis C, genotype 1, and 37 with genotype 4 with cirrhosis or recurrence after liver transplant who were treated with sofosbuvir, ledipasvir and ribavirin for 12 or 24 weeks, 72 patients [22%] had a serious adverse event and 17 died [5%], mainly from hepatic decompensation).
Issa D, Eghtesad B, Zein NN, Yerian L, Cruise M, Alkhouri N, Adams R, et al. (2016). Sofosbuvir and simeprevir for the treatment of recurrent hepatitis C with fibrosing cholestatic hepatitis after liver transplantation. Int J Organ Transplant Med. (Among 5 patients with recurrent hepatitis C and fibrosing cholestatic hepatitis after liver transplant who were treated with sofosbuvir and simeprevir for 24 weeks, 4 had an SVR with resolution of jaundice, and one developed hepatic decompensation and died).
Chuang WL, Chien RN, Peng CY, Chang TT, Lo GH, Sheen IS, Wang HY, et al. (2016). Ledipasvir/sofosbuvir fixed-dose combination tablet in Taiwanese patients with chronic genotype 1 hepatitis C virus. J Gastroenterol Hepatol. (Among 85 Chinese patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir for 12 weeks, 83 [98%] had an SVR, and none had a liver related adverse event).
Pillai AA, Wedd J, Norvell JP, Parekh S, Cheng N, Young N, Spivey JR, et al. (2016). Simeprevir and sofosbuvir (SMV-SOF) for 12 weeks for the treatment of chronic hepatitis C genotype 1 infection: a real world (transplant) hepatology practice experience. Am J Gastroenterol. (Among 170 patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir with or without ribavirin for 12 weeks in routine clinical practice, 133 [78%] had an SVR; adverse events were not discussed).
Abergel A, Asselah T, Metivier S, Kersey K, Jiang D, Mo H, Pang PS, et al. (2016). Ledipasvir-sofosbuvir in patients with hepatitis C virus genotype 5 infection: an open-label, multicentre, single-arm, phase 2 study. Lancet Infect Dis. (Among 41 patients with chronic hepatitis C, genotype 5, treated with sofosbuvir and ledispasvir for 12 weeks, 39 [95%] had an SVR, and there were no serious liver related adverse events).
Mandorfer M, Schwabl P, Steiner S, Scheiner B, Chromy D, Bucsics T, Stättermayer AF, et al. (2016). Interferon-free treatment with sofosbuvir/daclatasvir achieves sustained virologic response in 100% of HIV/HCV-coinfected patients with advanced liver disease. AIDS. (Among 31 patients with chronic hepatitis C with advanced fibrosis or cirrhosis and HIV coinfection who were treated with sofosbuvir and daclatasvir to 12 or 24 weeks, all had an SVR, and there were no discontinuations because of adverse events).
Brown RS, O'Leary JG, Reddy KR, Kuo A, Morelli GJ, Burton JR, Stravitz RT, et al. (2016). Hepatitis C Therapeutic Registry Research Network Study Group. Interferon-free therapy for genotype 1 hepatitis C in liver transplant recipients: Real-world experience from the hepatitis C therapeutic registry and research network. Liver Transpl. (Among 151 patients with recurrent hepatitis C after liver transplantation treated with sofosbuvir and simeprevir with or without ribavirin for 12 or 24 weeks, 133 [88%] had an SVR, and 8 [5%] developed hepatic decompensation and 3 patients died, all of whom had cirrhosis).
Lai CL, Wong VW, Yuen MF, Yang JC, Knox SJ, Mo H, Han LL, et al. (2016). Sofosbuvir plus ribavirin for the treatment of patients with chronic genotype 1 or 6 hepatitis C virus infection in Hong Kong. Aliment Pharmacol Ther. (Among 31 patients with chronic hepatitis C [genotype 1 or 4] treated with sofosbuvir and ribavirin for 12, 16 or 24 weeks, 30 [97%] had an SVR, and there were no serious adverse events and no mention of ALT elevations).
Sulkowski MS, Vargas HE, Di Bisceglie AM, Kuo A, Reddy KR, Lim JK, Morelli G, et al., HCV-TARGET Study Group. (2016). Effectiveness of simeprevir plus sofosbuvir, with or without ribavirin, in real-world patients with HCV genotype 1 infection. Gastroenterology. (Among 802 patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir with or without ribavirin for 12 weeks in clinical practices ["the real world"], 675 [84%] had an SVR, 44 [5.3%] had a serious adverse event, 10 [1.2%] hepatic decompensation and 2 [0.3%] died of liver failure).
Modi AA, Nazario H, Trotter JF, Gautam M, Weinstein J, Mantry P, Barnes M, et al. (2016). Safety and efficacy of simeprevir plus sofosbuvir with or without ribavirin in patients with decompensated genotype 1 hepatitis C cirrhosis. Liver Transpl. (Among 42 patients with chronic hepatitis C, genotype 1, and decompensated cirrhosis treated with sofosbuvir, simeprevir and [n=35] ribavirin for 12 weeks, 31 [74%] had an SVR, and none developed decompensation requiring hospitalization).
Fontana RJ, Brown RS, Moreno-Zamora A, Prieto M, Joshi S, Londoño MC, et al. (2016). Daclatasvir combined with sofosbuvir or simeprevir in liver transplant recipients with severe recurrent hepatitis C infection. Liver Transpl. (Among 97 liver transplant recipients treated with daclatasvir and either sofosbuvir or simeprevir with or without ribavirin for up to 24 weeks, 84 [87%] had an SVR, and 8 [8%] patients died, but none of the deaths were considered due to the antiviral therapy).
Poordad F, Schiff ER, Vierling JM, Landis C, Fontana RJ, Yang R, McPhee F, Hughes EA, Noviello S, Swenson ES. (2016). Daclatasvir with sofosbuvir and ribavirin for HCV infection with advanced cirrhosis or post-liver transplant recurrence. Hepatology. (Among 60 patients with advanced cirrhosis and 53 transplant recipients with chronic hepatitis C who were treated with daclatasvir, sofosbuvir and ribavirin for 12 weeks, SVR rates were 93% in Child-Pugh class A and B cirrhosis and 56% in class C, and 95% in transplant patients, and "there were no treatment related serious adverse events").
Dyson JK, Hutchinson J, Harrison L, Rotimi O, Tiniakos D, Foster GR, Aldersley MA, et al. (2016). Liver toxicity associated with sofosbuvir, an NS5A inhibitor and ribavirin use. J Hepatol. (74 year old man and 36 year old woman with HCV related cirrhosis developed worsening hepatic decompensation within a few weeks of starting sofosbuvir, an NS5A inhibitor and ribavirin [peak bilirubin 23.4 and 30.5 mg/dL, ALT 65 and 96 U/L, Alk P 202 and 398 U/L], resulting in death in one and emergency liver transplant in the other [Case 1]).
Marchan-Lopez A, Dominguez-Dominguez L, Kessler-Saiz P, Jarrin-Estupiñan ME. (2016). Liver failure in human immunodeficiency virus - hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy. J Hepatol. (Letter in response to Dyson [2016]: 49 year old man with chronic hepatitis C, cirrhosis [Child-Pugh class B] and HIV coinfection developed worsening hepatic decompensation 1 to 2 months after starting sofosbuvir and ledipasvir that worsened for two weeks after stopping [peak bilirubin 46.9 mg/dL, INR 3.17], and then resolved; he later tolerated reinitiation of antiretroviral drugs).
Dyson JK, McPherson S. (2016). Reply to "Liver failure in human immunodeficiency virus - Hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy". J Hepatol. (Letter in reply to March-Lopez [2016] reporting another case of hepatic decompensation during sofosbuvir, ledipasvir and ribavirin therapy of a patient hepatitis C, cirrhosis and HIV coinfection, arising within 6 weeks of starting treatment [bilirubin 12.6 mg/dL, protime 17 sec], and leading to successful, emergency liver transplantation).
Welker MW, Luhne S, Lange CM, Vermehren J, Farnik H, Herrmann E, Welzel T, et al. (2016). Lactic acidosis in patients with hepatitis C virus cirrhosis and combined ribavirin/ sofosbuvir treatment. J Hepatol. (Among 35 patients with chronic hepatitis C and advanced fibrosis or cirrhosis treated with sofosbuvir based regimens, 12 [34%] had a serious adverse event and 5 [14%] developed lactic acidosis, largely in those with Child-Pugh class B or C cirrhosis and in the context of hepatic decompensation, 2 of whom died).
Hoofnagle JH. (2016). Hepatic decompensation during direct-acting antiviral therapy of chronic hepatitis C. J Hepatol. (Editorial in response to Welker [2016] discussing the occurrence of unexplained hepatic decompensation during antiviral therapy of hepatitis C and whether these episodes are coincidental, caused by hepatoxicity of the antiviral drugs, or are the paradoxical result of sudden eradication of the chronic viral infection).
Lawitz E, Reau N, Hinestrosa F, Rabinovitz M, Schiff E, Sheikh A, Younes Z, et al. (2016). Efficacy of sofosbuvir, velpatasvir, and GS-9857 in patients with genotype 1 hepatitis C virus infection in an open-label, phase 2 trial. Gastroenterology. (Among 197 patients with chronic hepatitis C, genotype 1, treated with sofosbuvir-velpatsavir-voxilaprevir for 6, 8 or 12 weeks, SVR rates were 100% with the 12 week regimen regardless of previous therapy or cirrhosis, while side effects were generally mild, but one patient with cirrhosis discontinued therapy early because of ALT levels above 5 times ULN and mild bilirubin increases, which resolved within 4 weeks of stopping).
Gane EJ, Kowdley KV, Pound D, Stedman CA, Davis M, Etzkorn K, Gordon SC, et al. (2016). Efficacy of sofosbuvir, velpatasvir, and GS-9857 in patients with hepatitis C virus genotype 2, 3, 4, or 6 infections in an open-label, phase 2 trial. Gastroenterology. (Among 128 patients with chronic hepatitis C, genotypes 2, 3, 4 or 6, who were treated with sofosbuvir-velpatsavir-voxilaprevir or 6, 8 or 12 weeks, SVR rates were 97-100% with 12 weeks of therapy and adverse events were generally mild; no patient developed clinically apparent liver injury, hepatic decompensation or a late rise in serum ALT levels).
Gane EJ, Schwabe C, Hyland RH, Yang Y, Svarovskaia E, Stamm LM, Brainard DM, et al. (2016). Efficacy of the combination of sofosbuvir, velpatasvir, and the NS3/4A protease inhibitor GS-9857 in treatment-naïve or previously treated patients with hepatitis C virus genotype 1 or 3 infections. Gastroenterology. (Among 161 patients with chronic hepatitis C treated with sofosbuvir, velpatasvir and voxilaprevir for 4, 6 or 8 weeks, SVR rates of 89-100% were obtained only with the 8-week courses, and no patient developed hepatic decompensation or clinically apparent liver injury with jaundice).
Lawitz E, Poordad F, Hyland RH, Wang J, Liu L, Dvory-Sobol H, Brainard DM, et al. (2016). Ledipasvir/sofosbuvir-based treatment of patients with chronic genotype-1 HCV infection and cirrhosis: results from two Phase II studies. Antivir Ther. (Among 146 patients with cirrhosis and chronic hepatitis C, genotype 1, treated with 8 weeks of sofosbuvir and ledipasvir combined with ribavirin, vedroprevir or GS9669, the SVR rate ranged from 82-95% and no liver related adverse events were reported).
Ingiliz P, Christensen S, Kimhofer T, Hueppe D, Lutz T, Schewe K, Busch H, et al. (2016). Sofosbuvir and ledipasvir for 8 weeks for the treatment of chronic hepatitis C virus (HCV) infection in HCV-monoinfected and HIV-HCV-coinfected individuals: results from the German Hepatitis C Cohort (GECCO-01). Clin Infect Dis. (Among 193 patients with chronic hepatitis C treated with sofosbuvir and ledipasvir for 8 weeks, 186 [94%] had an SVR; serious adverse events were not reported).
Kwok RM, Ahn J, Schiano TD, Te HS, Potosky DR, Tierney A, Satoskar R, et al. (2016). Sofosbuvir plus ledispasvir for recurrent hepatitis C in liver transplant recipients. Liver Transpl. (Among 204 patients with chronic hepatitis C after liver transplantation who were treated with sofosbuvir and ledipasvir for 8 or 12 weeks, the SVR rate was 96% and "no significant serious adverse events were documented" although 4 patients died, and one suffered graft rejection and one stopped therapy early because of a rise in both ALT and bilirubin levels).
Benítez-Gutiérrez L, de Mendoza C, Baños I, Duca A, Arias A, Treviño A, Requena S, et al. (2016). Drug-induced lung injury in a liver transplant patient treated With sofosbuvir. Transplant Proc. (Among 24 liver transplant recipients with chronic hepatitis C treated with sofosbuvir containing antiviral regimens, 23 [95%] achieved an SVR, but one developed severe respiratory failure [suspected drug induced lung injury] 10 days after starting therapy, which was successfully treated with prednisone and she was later was successfully treated with 24 weeks of daclatasvir and simeprevir and achieved an SVR).
Alonso S, Riveiro-Barciela M, Fernandez I, Rincón D, Real Y, Llerena S, Gea F, et al. (2017). Effectiveness and safety of sofosbuvir-based regimens plus an NS5A inhibitor for patients with HCV genotype 3 infection and cirrhosis. results of a multicenter real-life cohort. J Viral Hepat. (Among 208 cirrhotic patients with chronic hepatitis C, genotype 3, treated with sofosbuvir and either daclatasvir or lepidasvir with or without ribavirin, the overall SVR rate was 94% and 7 patients developed hepatic decompensation, 3 of whom died).
Pol S, Bourliere M, Lucier S, Hezode C, Dorival C, Larrey D, Bronowicki JP, et al., ANRS/AFEF HEPATHER study group. (2017). Safety and efficacy of daclatasvir-sofosbuvir in HCV genotype 1-mono-infected patients. J Hepatol. (Among 768 patients with chronic hepatitis C treated in community practice with sofosbuvir and daclatasvir, the overall SVR rate was 95% and was similar for 12 and 24 weeks of treatment, with or without ribavirin; there were 5 deaths, 2 from end stage liver disease that were considered unrelated to therapy).
Welzel TM, Petersen J, Herzer K, Ferenci P, Gschwantler M, Wedemeyer H, Berg T, et al. (2016). Daclatasvir plus sofosbuvir, with or without ribavirin, achieved high sustained virological response rates in patients with HCV infection and advanced liver disease in a real-world cohort. Gut. (Among 460 patients with chronic hepatitis C treated with sofosbuvir and daclatasvir in a European compassionate use program between 2014 and 2015, the overall SVR rate was 91%, while 94 [19%] had a serious adverse event and 28 died [6%], most commonly from hepatic failure; there were no reports of reactivation of hepatitis B).
Sperl J, Horvath G, Halota W, Ruiz-Tapiador JA, Streinu-Cercel A, Jancoriene L, Werling K, et al. (2016). Efficacy and safety of elbasvir/grazoprevir and sofosbuvir/pegylated interferon/ribavirin: A phase III randomized controlled trial. J Hepatol. (Among 257 patients with chronic hepatitis C, genotypes 1 and 4, SVR rates were 99% with 12 weeks of elbasvir and grazoprevir and 90.5% with 12 weeks of sofosbuvir, peginterferon and ribavirin; adverse events were more frequent in the interferon treated subjects, but there were no deaths and no liver related serious adverse events or late ALT elevations).
Feld JJ, Maan R, Zeuzem S, Kuo A, Nelson DR, Di Bisceglie AM, Manns MP, et al. (2016). Effectiveness and safety of sofosbuvir-based regimens for chronic HCV genotype 3 infection: results of the HCV-TARGET Study. Clin Infect Dis. (Among 178 patients with chronic hepatitis C, genotype 3, treated with sofosbuvir and ribavirin, the overall response rate was 60% and 11 patients had a decompensation event, arising 0.1 to 24 weeks after starting, all with a previous history of decompensation).
Coilly A, Fougerou-Leurent C, de Ledinghen V, Houssel-Debry P, Duvoux C, Di Martino V, Radenne S, et al. (2016). ANRS C023 CUPILT study group. Multicentre experience using daclatasvir and sofosbuvir to treat hepatitis C recurrence - The ANRS CUPILT study. J Hepatol. (Among 137 patients with recurrent hepatitis C after liver transplantation treated in a compassionate use program with sofosbuvir and daclatasvir between 2013 and 2015, the overall SVR rate was 96% and was no higher with addition of ribavirin; the serious adverse event rate was 18%, 2 patients had an episode of graft rejection, and 2 died [1.5%], one of hyperosmolar coma arising within a week of starting therapy and one of hepatocellular carcinoma).
Bourlière M, Gordon SC, Flamm SL, Cooper CL, Ramji A, Tong M, Ravendhran N, et al., POLARIS-1 and POLARIS-4 Investigators. (2017). Sofosbuvir, velpatasvir, and voxilaprevir for previously treated HCV infection. N Engl J Med. (Among 708 patients with chronic hepatitis C and previous therapy direct acting antivirals, SVR rates were 98% for sofosbuvir-velpatasvir-voxilaprevir vs 91% with sofosbuvir-velpatasvir alone and adverse events more frequent with triple therapy included headache, diarrhea and nausea; only one patient had an ALT elevation above 5 times ULN).
Jacobson IM, Lawitz E, Gane EJ, Willems BE, Ruane PJ, Nahass RG, Borgia SM, et al. (2017). Efficacy of 8 weeks of sofosbuvir, velpatasvir, and voxilaprevir in patients with chronic HCV infection: 2 phase 3 randomized trials. Gastroenterology. (Among 828 treatment-naive patients with chronic hepatitis C, genotypes 1 through 6, who were treated with 8 weeks of sofosbuvir-velpatasvir-voxilaprevir or 12 weeks of sofosbuvir-velpatasvir alone, SVR rates were 95-98%, and adverse events were generally mild, one patient developed transient elevations of ALT more than 5 times ULN, but there were no serious hepatic adverse events and no early discontinuations for liver related test abnormalities).
Lawitz E, Poordad F, Wells J, Hyland RH, Yang Y, Dvory-Sobol H, Stamm LM, et al. (2017). Sofosbuvir-velpatasvir-voxilaprevir with or without ribavirin in direct-acting antiviral-experienced patients with genotype 1 hepatitis C virus. Hepatology. (Among 49 patients with chronic hepatitis C, genotype 1, previously treated with direct acting antiviral agents, who were treated with sofosbuvir-velpatasvir-voxilaprevir, with or without ribavirin for 12 weeks, all except 1 had an SVR and adverse events were generally mild, one patient developed transient elevations of ALT more than 5 times ULN, but there were no serious hepatic adverse events and no early discontinuations for liver related test abnormalities).
Gane EJ, Shiffman ML, Etzkorn K, Morelli G, Stedman C, Davis MN, Hinestrosa F, et al. (2017). GS-US-342-1553 Investigators. Sofosbuvir-velpatasvir with ribavirin for 24 weeks in HCV patients previously treated with a direct-acting antiviral regimen. Hepatology. (Among 69 patients with chronic hepatitis C who had failed to respond to a course of direct acting antiviral therapy and were treated with a 24-week course of sofosbuvir-velpatasvir and ribavirin, the SVR rate was 91% and adverse events were largely due to ribavirin, and there were no ALT elevations after the initial decrease).
Liu CJ, Chuang WL, Sheen IS, Wang HY, Chen CY, Tseng KC, Chang TT, et al. (2018). Efficacy of ledipasvir and sofosbuvir treatment of HCV infection in patients coinfected with HBV. Gastroenterology. (Among 111 Taiwanese patients with chronic hepatitis C and HBsAg in serum who were treated with sofosbuvir and ledipasvir for 12 weeks, all achieved an SVR [100%] and 31 of 37 [87%] without detectable HBV DNA initially developed low levels during therapy, while 39 of 74 [53%] with detectable HBV DNA initially had a rise in concentration; only 5 of the 70 patients with HBV reactivation had modest ALT elevations of whom 3 received anti-HBV therapy).
Bersoff-Matcha SJ, Cao K, Jason M, Ajao A, Jones SC, Meyer T, Brinker A. (2017). Hepatitis B virus reactivation associated with direct-acting antiviral therapy for chronic hepatitis C virus: a review of cases reported to the U.S. Food and Drug Administration adverse event reporting system. Ann Intern Med. (FDA summary of 29 reports of HBV reactivation among patients with chronic hepatitis C being treated with DAAs, presenting 14-196 days after starting therapy with various DAA regimens, 3 resulting in death, 19 from Japan, 5 from the US, many treated after a delay in identifying the cause of sudden worsening of liver disease).
Mahale P, Glenn JS, O'Brien TR. (2017). Hepatitis B virus reactivation associated with direct-acting antiviral therapy for chronic hepatitis C virus. Ann Intern Med. (Letter in response to Bersoff-Matcha [2017] suggesting that some cases of sudden worsening of liver disease in HBsAg positive patients might be due to superinfections with hepatitis D [Delta] virus).
Bersoff-Matcha SJ, Cao K, Jason M, Jones SC, Brinker A. (2017). Hepatitis B virus reactivation associated with direct-acting antiviral therapy for chronic hepatitis C virus. Ann Intern Med. (Reply to the letter to the editor by Mahale [2017] by the authors).
Serper M, Forde KA, Kaplan DE. (2018). Rare clinically significant hepatic events and hepatitis B reactivation occur more frequently following rather than during direct-acting antiviral therapy for chronic hepatitis C: Data from a national US cohort. J Viral Hepat. (Analysis of the large VA Medical system database of 17,400 veterans with chronic hepaittis C as well as anti-HBc who received oral DAA therapy, identified only 2 cases of HBV reactivation with serum ALT elevations above 300 U/L among 97 HBsAg positive patients).
Aggeletopoulou I, Konstantakis C, Manolakopoulos S, Triantos C. (2017). Risk of hepatitis B reactivation in patients treated with direct-acting antivirals for hepatitis C. World J Gastroenterol. (Review of the literature on reactivation of HBV during antiviral therapy of chronic hepatitis C summarizing 7 cases in the literature).
Calvaruso V, Ferraro D, Licata A, Bavetta MG, Petta S, Bronte F, Colomba G, et al. (2018). HBV reactivation in patients with HCV/HBV cirrhosis on treatment with direct-acting antivirals. J Viral Hepat. (Among 104 patients with cirrhosis and chronic hepatitis C who were treated with DAAs, reactivation of HBV occurred in 3 of 4 HBsAg positive patients not on anti-HBV therapy, but none developed ALT elevations or clinically apparent acute liver injury).
Loggi E, Gitto S, Galli S, Minichiello M, Conti F, Grandini E, Scuteri A, et al. (2017). Hepatitis B virus reactivation among hepatitis C patients treated with direct-acting antiviral therapies in routine clinical practice. J Clin Virol. (Among 137 Italian adults with chronic hepatitis C treated with DAAs during a one year period, reactivation [without ALT elevations] occurred in 1 of 2 subjects with HBsAg, but in none of 42 with anti-HBc without HBsAg).
Huang R, Yan X, Xia J, Wang J, Wu C. (2017). Letter: hepatitis B virus reactivation in patients with chronic hepatitis C during direct-acting anti-viral therapy. Aliment Pharmacol Ther. (Letter in response to Londono [2017] pointing out the differing definitions of HBV reactivation and "occult" hepatitis B used in the literature).
Londoño MC, Carrión JA, Forns X. (2017). Letter: hepatitis B reactivation in patients with chronic hepatitis C during direct-acting antiviral therapy-authors' reply. Aliment Pharmacol Ther. (Reply to the letter to the editor by Huang [2017] by the authors).
Kawagishi N, Suda G, Onozawa M, Kimura M, Maehara O, Ito J, Nakai M, et al. (2017). Hepatitis B virus reactivation during hepatitis C direct-acting antiviral therapy in patients with previous HBV infection. J Hepatol. (Letter describing course of 5 of 84 patients with chronic hepatitis C and serologic evidence of previous HBV infection [anti-HBc without HBsAg] developed evidence of HBV reactivation during various DAA regimens that was not accompanied by ALT elevations, but was persistent after DAA treatment in two patients).
Fabbri G, Mastrorosa I, Vergori A, Mazzotta V, Pinnetti C, Grisetti S, Zaccarelli M, et al. (2017). Reactivation of occult HBV infection in an HIV/HCV co-infected patient successfully treated with sofosbuvir/ledipasvir: a case report and review of the literature. BMC Infect Dis. (54 year old woman with HCV/HIV coinfection and anti-HBc without HBsAg in serum developed reactivation of hepatitis B [HBsAg and HBeAg positive] with acute hepatitis and jaundice 4 weeks after stopping DAA therapy [bilirubin 7.1 mg/dL< ALT 435 U/L, HBV DNA 6.1 log IU/mL], jaundice and aminotransferase elevations resolving within a month of starting entecavir).
Belperio PS, Shahoumian TA, Mole LA, Backus LI. (2017). Evaluation of hepatitis B reactivation among 62,920 veterans treated with oral hepatitis C antivirals. Hepatology. (Analysis of VA Medical Database of 62,920 veterans with chronic hepatitis C treated with oral DAAs of whom 9 had evidence of HBV reactivation, 8 in patients with HBsAg and 1 with anti-HBc without HBsAg in serum, but only 3 patients had ALT elevations above twice ULN).
Yeh ML, Huang CF, Hsieh MH, Ko YM, Chen KY, Liu TW, Lin YH, et al. (2017). Reactivation of hepatitis B in patients of chronic hepatitis C with hepatitis B virus infection treated with direct acting antivirals. J Gastroenterol Hepatol. (Among 64 patients with chronic hepatitis C and serologic evidence of ongoing or previous HBV infection who were treated with various DAA regimens, 4 of 7 HBsAg positive [57%], but none of 57 anti-HBc positive, HBsAg negative subjects developed HBV reactivation but all cases were subclinical, ALT elevations occurring in only one).
Londoño MC, Lens S, Mariño Z, Bonacci M, Ariza X, Broquetas T, Pla A, et al. (2017). Hepatitis B reactivation in patients with chronic hepatitis C undergoing anti-viral therapy with an interferon-free regimen. Aliment Pharmacol Ther. (Among 352 patients with chronic hepatitis C receiving DAA treatment, 5 of 10 [50%] with concurrent HBsAg and 1 of 64 with anti-HBc without HBsAg developed a 1 log IU/mL increase in HBV DNA levels, but elevations were modest and none developed ALT elevations or clinically apparent liver injury).
Kawagishi N, Suda G, Onozawa M, Kimura M, Maehara O, Ohara M, Izumi T, et al. (2017). Comparing the risk of hepatitis B virus reactivation between direct-acting antiviral therapies and interferon-based therapies for hepatitis C. J Viral Hepat. (Among 151 patients with chronic hepatitis C undergoing antiviral therapy, reactivation of HBV occurred in 1 of 4 patients with HBsAg in serum, and 5 of 151 with anti-HBc without HBsAg, but peak HBV DNA levels were low and all cases were without ALT elevations or symptoms and all 6 occurred in 79 patients receiving oral DAAs [8%] and none in the 72 who received interferon-based therapies [0%]).
Mücke VT, Mücke MM, Peiffer KH, Weiler N, Welzel TM, Sarrazin C, Zeuzem S, et al. (2017). No evidence of hepatitis B virus reactivation in patients with resolved infection treated with direct-acting antivirals for hepatitis C in a large real-world cohort. Aliment Pharmacol Ther. (Among 848 patients with chronic hepatitis C treated in the "real world" with DAAs, 5 of 9 patients with HBsAg developed HBV reactivation [3 ultimately requiring anti-HBV therapy] and 8 of 263 patients with anti-HBc without HBsAg had low, but detectable levels of HBV DNA during therapy, but without ALT elevations).
(2016). In brief: Hepatitis B reactivation with direct-acting antiviral drugs for hepatitis C. Med Lett Drugs Ther. (Brief summary of the FDA warning letter concerning HBV reactivation caused by DAA therapies of hepatitis C).
Sulkowski MS, Chuang WL, Kao JH, Yang JC, Gao B, Brainard DM, Han KH, et al. (2016). No evidence of reactivation of hepatitis B virus among patients treated with ledipasvir-sofosbuvir for hepatitis C virus infection. Clin Infect Dis. (Among 173 Taiwanese and Korean patients with chronic hepatitis C treated with 12 weeks of sofosbuvir and ledipasvir, the SVR rate was 98% and retrospective testing of follow up samples demonstrated anti-HBc without HBsAg in 103 [60%], two of whom had low and unquantifiable levels of HBV DNA, but none had acute ALT elevations or clinical evidence of HBV reactivation).
Wang C, Ji D, Chen J, Shao Q, Li B, Liu J, Wu V, et al. (2017). Hepatitis due to Reactivation of hepatitis B virus in endemic areas among patients with hepatitis C treated with direct-acting antiviral agents. Clin Gastroenterol Hepatol. (Among 327 Chinese patients with chronic hepatitis C treated with various DAA regimens, the overall SVR rate was 99% and 3 of 10 patients [30%] with HBsAg in serum developed clinically apparent HBV reactivation [and one died], compared to one of 124 patients [1%] with anti-HBc without HBsAg and none of 193 without anti-HBc).
Hayashi K, Ishigami M, Ishizu Y, Kuzuya T, Honda T, Nishimura D, Goto H, et al. (2016). A case of acute hepatitis B in a chronic hepatitis C patient after daclatasvir and asunaprevir combination therapy: hepatitis B virus reactivation or acute self-limited hepatitis?. Clin J Gastroenterol. (83 year old woman with chronic hepatitis C and no HBsAg in serum was treated with daclatasvir and asunaprevir and achieved an SVR, but presented 5 months later with an acute reactivation of hepatitis B).
Takayama H, Sato T, Ikeda F, Fujiki S. (2016). Reactivation of hepatitis B virus during interferon-free therapy with daclatasvir and asunaprevir in patient with hepatitis B virus/hepatitis C virus co-infection. Hepatol Res. (69 year old Japanese man with chronic hepatitis C and HBsAg in serum with low levels of HBV DNA developed reactivation of HBV 5 to 6 weeks after starting daclatasvir and asunaprevir with rise in ALT levels to 237 U/L, HBV DNA 10 million IU/mL and response to withdrawal of HCV therapy and addition of entecavir).
Kutala BK, Mouri F, Castelnau C, Bouton V, Giuily N, Boyer N, Asselah T, et al. (2017). Efficacy and safety of sofosbuvir-based therapies in patients with advanced liver disease in a real-life cohort. Hepat Med. (Among 374 patients with chronic hepatitis C and cirrhosis or advanced fibrosis who were treated with sofosbuvir, SVR rates were 82% with ribavirin, 97% with daclatasvir and 79% with simeprevir, and hepatic decompensation occurred in only one patient who received ribavirin; no details provided).
Navarro J, Laguno M, Vilchez HH, Guardiola JM, Carrion JA, Force L, Cairó M, et al., Catalano-Balear Study Group. (2017). Efficacy and safety of direct antiviral agents in a cohort of cirrhotic HCV/HIV-coinfected patients. J Antimicrob Chemother. (Among 170 cirrhotic patients with chronic hepatitis C and HIV coinfection treated with DAAs at 13 Spanish hospitals, the overall SVR rate was 93% and 4 patients [2.4%] developed hepatic decompensation during therapy).
Medeiros T, Salviato CM, do Rosário NF, Saraiva GDN, Esberard EBC, Almeida JR, Xavier AR, et al. (2017). Adverse effects of direct acting antiviral-based regimens in chronic hepatitis C patients: a Brazilian experience. Int J Clin Pharm. (Among 102 Brazilian patients with chronic hepatitis C treated with DAAs for 12 or 24 weeks, 100% had an SVR and adverse events were usually mild; no mention of ALT elevations or hepatic decompensation).
Wyles D, Bräu N, Kottilil S, Daar ES, Ruane P, Workowski K, Luetkemeyer A, et al. (2017). ASTRAL-5 Investigators. Sofosbuvir and velpatasvir for the treatment of hepatitis C virus in patients coinfected with human immunodeficiency virus type 1: an open-label, phase 3 study. Clin Infect Dis. (Among 106 patients with chronic hepatitis C and HIV coinfection treated with sofosbuvir and velpatasvir for 12 weeks, the SVR rate was 95% and serious adverse events occurred in only 2 patients, one of whom with cirrhosis had worsening of ALT and bilirubin levels and stopped therapy early but achieved an SVR).
Calleja JL, Crespo J, Rincón D, Ruiz-Antorán B, Fernandez I, Perelló C, Gea F, et al. (2017). Spanish Group for the Study of the Use of Direct-acting Drugs Hepatitis C Collaborating Group. Effectiveness, safety and clinical outcomes of direct-acting antiviral therapy in HCV genotype 1 infection: Results from a Spanish real-world cohort. J Hepatol. (Among 1758 patients with chronic hepatitis C treated with sofosbuvir and ledipasvir with or without ribavirin at 35 Spanish centers, the SVR rate was 96%, and 97 patients had a serious adverse event and 16 hepatic decompensation [1%], all of whom had cirrhosis and 3 of whom died of liver failure).
Suda KJ, Halbur DJ, Hunkler RJ, Matusiak LM, Schumock GT. (2017). Spending on hepatitis C antivirals in the United States, 2009-2015. Pharmacotherapy. (Analysis of expenditures for therapy of hepatitis C in the US between 2009 and 2015 showed a rise from $77 million in 2009 to $1 billion in 2011 and $18 billion in 2015, the major expenditures being for sofosbuvir).
Tamori A, Abiru S, Enomoto H, Kioka K, Korenaga M, Tani J, Enomoto M, et al. (2018). Low incidence of hepatitis B virus reactivation and subsequent hepatitis in patients with chronic hepatitis C receiving direct-acting antiviral therapy. J Viral Hepat. (Among patients with chronic hepatitis C treated with DAAs, HBV reactivation occurred in 3 of 22 patients [14%] with concurrent HBsAg [and not on anti-HBV therapy] and in 1 of 765 [<1%] with resolved hepatitis B, but none of the affected patients had ALT elevations or clinically apparent acute liver injury).
Butt AA, Yan P, Shaikh OS, Abou-Samra AB. (2018). Hepatitis B reactivation and outcomes in persons treated with directly acting antiviral agents against hepatitis C virus: results from ERCHIVES. Aliment Pharmacol Ther. (Among patients with chronic hepatitis C treated in the VA Medical system, 9 of 377 [2%] with HBsAg receiving DAAs and 37 of 209 [18%] receiving peginterferon and ribavirin developed HBV reactivation).
Buggisch P, Vermehren J, Mauss S, Günther R, Schott E, Pathil A, Boeker K, et al. (2018). Real-world effectiveness of 8-week treatment with ledipasvir/sofosbuvir in chronic hepatitis C. J Hepatol. (Among 2,404 Germans with chronic hepatitis C treated with sofosbuvir and ledipasvir in community practice, SVR rates were similar with 8 weeks [85.1%] as 12 weeks [85.5%], but serious adverse events were less common with 8 weeks [1.7% vs 2.8%]).
Pol S, Bourliere M, Lucier S, Hezode C, Dorival C, Larrey D, Bronowicki JP, et al., ANRS/AFEF HEPATHER study group. (2017). Safety and efficacy of daclatasvir-sofosbuvir in HCV genotype 1-mono-infected patients. J Hepatol. (Among 798 patients with chronic hepatitis C, genotype 1, [80% with cirrhosis] treated with sofosbuvir and daclatasvir with or without ribavirin for 12 or 24 weeks, the overall SVR rate was 95%, cirrhotic patients having a higher SVR rate with 24 than 12 weeks [96% vs 92%]; two patients with cirrhosis died of end-stage liver disease at 11 and 24 weeks of treatment).
Modi AA, Nazario HE, Gonzales GR, Gonzalez SA. (2018). Safety and efficacy of ledipasvir/sofosbuvir with or without ribavirin in hepatitis C genotype 1 patients including those with decompensated cirrhosis who failed prior treatment with simeprevir/sofosbuvir. Aliment Pharmacol Ther. (Among 30 patients with chronic hepatitis C [62% with decompensated cirrhosis] who had failed to respond to sofosbuvir and simeprevir who were re-treated with sofosbuvir and ledipasvir with or without ribavirin for 12 or 24 weeks, the overall SVR rate was 90% and hospitalization with serious adverse events occurred in 2 patients with Child’s B cirrhosis [one variceal bleed and one for abdominal pain], but both recovered and did not stop therapy).
Sanai FM, Altraif IH, Alswat K, AlZanbagi A, Babatin MA, AlMousa A, Almutairi NH, et al. (2018). Real life efficacy of ledipasvir/sofosbuvir in hepatitis C genotype 4-infected patients with advanced liver fibrosis and decompensated cirrhosis. J Infect. (Among 213 Saudi Arabian patients with chronic hepatitis C, genotype 4, and advanced fibrosis [n=30] or compensated [n=135] or decompensated [n=48] cirrhosis, the overall SVR rate was 92.5% and was similar with or without ribavirin [ 92.6% vs 90.9%] and regardless of fibrosis stage [90% to 93%]; while severe adverse events arose in 9 patients, 8 developed or had worsening decompensation, and 3 died).
Hézode C, Lebray P, De Ledinghen V, Zoulim F, Di Martino V, Boyer N, Larrey D, et al. (2017). Daclatasvir plus sofosbuvir, with or without ribavirin, for hepatitis C virus genotype 3 in a French early access programme. Liver Int. (Among 333 adults with chronic hepatitis C, genotype 3, [cirrhosis in 77%] treated with sofosbuvir and daclatasvir for 24 weeks, the overall SVR rate was 89%, and was 88% in those with and 98% in those without cirrhosis, while the adverse event rate was 37%, serious adverse event rate 14%, 3 patients developed decompensation during treatment and one died of liver failure).
Saxena V, Khungar V, Verna EC, Levitsky J, Brown RS, Hassan MA, Sulkowski MS, et al. (2017). Safety and efficacy of current direct-acting antiviral regimens in kidney and liver transplant recipients with hepatitis C: Results from the HCV-TARGET study. Hepatology. (Among 412 patients with liver or kidney transplants or both and chronic hepatitis C treated with direct acting antiviral agents with or without ribavirin in a prospective observational study, the SVR rate was 96% with sofosbuvir and ledipasvir and somewhat lower with sofosbuvir and daclatasvir and Viekira Pak; serious adverse events occurred in 10% including hepatic encephalopathy in 2 patients).
El-Khayat H, Fouad Y, Mohamed HI, El-Amin H, Kamal EM, Maher M, Risk A. (2018). Sofosbuvir plus daclatasvir with or without ribavirin in 551 patients with hepatitis C-related cirrhosis, genotype 4. Aliment Pharmacol Ther. (Among 551 Egyptian adults with chronic hepatitis C, genotype 4, with cirrhosis treated with sofosbuvir and daclatasvir with ribavirin for 12 weeks and without ribavirin for 24 weeks, the SVR rate was 92%, and serious adverse events arose mostly in those with decompensated cirrhosis which included hepatic encephalopathy and liver cancer).
Kwo P, Fried MW, Reddy KR, Soldevila-Pico C, Khemichian S, Darling J, Zamor PJ, et al. (2018). Daclatasvir and sofosbuvir treatment of decompensated liver disease or post-liver transplant hepatitis C virus recurrence in patients with advanced liver disease/cirrhosis in a real-world cohort. Hepatol Commun. (Among 77 patients with chronic hepatitis C with decompensated cirrhosis [n=14] or recurrent hepatitis C after liver transplant treated with sofosbuvir and daclatasvir with or without ribavirin for 24 weeks, the SVR rate was 62% for those with decompensated cirrhosis and 90% with recurrence after transplantation; adverse events were reported in 90% of patients which were serious in 39%, leading to discontinuation of therapy in 13% and resulting in death in 6 [4 were liver related]).
Gaeta GB, Aghemo A, Menzaghi B, D'Offizi G, Giorgini A, Hasson H, Brancaccio G, et al., STIly Study Group. (2018). Effectiveness and safety of simeprevir-based regimens for hepatitis C in Italy: The STIly observational study. Medicine (Baltimore). (Among 342 Italian patients with chronic hepatitis C [genotypes 1 and 4] treated with 12 weeks of sofosbuvir and simeprevir with or without ribavirin, the overall SVR rate was 95% while serious adverse events arose in 1.2%, but all resolved without need for drug discontinuations; no mention of liver injury, hepatitis or ALT elevations).
Miotto N, Mendes LC, Zanaga LP, Lazarini MSK, Goncales ESL, Pedro MN, Goncales FL, Stucchi RSB, et al. (2018). All-oral direct antiviral treatment for hepatitis C chronic infection in a real-life cohort: The role of cirrhosis and comorbidities in treatment response. PLoS One. (Among 527 Brazilian patients with chronic hepatitis C treated with interferon free regimens [including sofosbuvir, daclatasvir, ribavirin and simeprevir] between 2015 and 2018, the overall SVR rate was 91% and 22 of 272 patients [8%] with cirrhosis had decompensation during therapy).
Bourlière M, Gordon SC, Schiff ER, Tran TT, Ravendhran N, Landis CS, Hyland RH, et al. (2018). Deferred treatment with sofosbuvir-velpatasvir-voxilaprevir for patients with chronic hepatitis C virus who were previously treated with an NS5A inhibitor: an open-label substudy of POLARIS-1. Lancet Gastroenterol Hepatol. (Among 155 patients with chronic hepatitis C and compensated cirrhosis who had failed to respond to previous interferon-based regimens and who were treated with sofosbuvir and ledipasvir, either with ribavirin for 12 weeks or with placebo for 24 weeks, the SVR rate was similar in the two groups [12 weeks 96% and 24 weeks 97%] and there were no episodes of hepatic decompensation).
Yanny BT, Latt NL, Saab S, Han S, Choi G, Kramer J, Sahota AK. (2018). Risk of hepatitis B virus reactivation among patients treated with ledipasvir-sofosbuvir for hepatitis C virus infection. J Clin Gastroenterol. (Among 1980 patients with chronic hepatitis C treated with sofosbuvir and lepidasvir in 2015-2016 in the Kaiser Permanente Medical System, 155 were HBsAg positive [98 on therapy of HBV, 57 not] and 127 had anti-HBc without HBsAg, but none developed reactivation of hepatitis B during therapy).
Murray KF, Balistreri WF, Bansal S, Whitworth S, Evans HM, Gonzalez-Peralta RP, Wen J, et al. (2018). Safety and efficacy of ledipasvir-sofosbuvir with or without ribavirin for chronic hepatitis C in children ages 6-11. Hepatology. (Among 92 children ages 6 to 12 with chronic hepatitis C treated with sofosbuvir and ledipasvir [200 mg and 45 mg] once daily with or without ribavirin for 12 or 24 weeks, the SVR rate was 99% overall and there were no hepatic related adverse events).
Shiha G, Soliman R, ElBasiony M, Hassan AA, Mikhail NNH. (2018). Sofosbuvir plus daclatasvir with or without ribavirin for treatment of chronic HCV genotype 4 patients: real-life experience. Hepatol Int. (Among 1168 Egyptian adults with chronic hepatitis C, genotype 4, treated with sofosbuvir and daclatasvir with or without ribavirin for 12 or 24 weeks, the SVR rate was 97% and there were no serious adverse events and only one patient discontinued therapy early for side effects).
Miotto N, Mendes LC, Zanaga LP, Lazarini MSK, Goncales ESL, Pedro MN, Goncales FL, Stucchi RSB, et al. (2018). All-oral direct antiviral treatment for hepatitis C chronic infection in a real-life cohort: The role of cirrhosis and comorbidities in treatment response. PLoS One. (Among 527 Brazilian patients with chronic hepatitis C treated with interferon free regimens [including sofosbuvir, daclatasvir, ribavirin and simpeprevir] between 2015 and 2018, the overall SVR rate was 91% and 22 of 272 patients [8%] with cirrhosis had decompensation during therapy).
Cheng PN, Chiu YC, Chien SC, Chiu HC. (2019). Real-world effectiveness and safety of sofosbuvir plus daclatasvir with or without ribavirin for genotype 2 chronic hepatitis C in Taiwan. J Formos Med Assoc. (Among 32 Taiwanese adults with chronic hepatitis C, genotype 2, [50% with cirrhosis, decompensated in 19%] treated with sofosbuvir and daclatasvir for 12 weeks, the SVR rate was 100%; 1 patient had a transient ALT elevation above 5 times ULN, and severe adverse events included a death from heart failure in one patient and transient hepatic encephalopathy in another).
Poordad F, Shiffman ML, Ghesquiere W, Wong A, Huhn GD, Wong F, Ramji A, et al. (2019). ALLY-3C study team. Daclatasvir and sofosbuvir with ribavirin for 24 weeks in chronic hepatitis C genotype-3-infected patients with cirrhosis: a Phase III study (ALLY-3C). Antivir Ther. (Among 78 patients with chronic hepatitis C, genotype 3, with compensated cirrhosis treated with sofosbuvir and daclatasvir without ribavirin for 24 weeks, the SVR rate was 87% and there were no deaths, but 8 serious adverse events, but none were liver related).
Wei L, Lim SG, Xie Q, Văn KN, Piratvisuth T, Huang Y, Wu S, Xu M, et al. (2019). Sofosbuvir-velpatasvir for treatment of chronic hepatitis C virus infection in Asia: a single-arm, open-label, phase 3 trial. Lancet Gastroenterol Hepatol. (Among 375 patients with chronic hepatitis C treated with sofosbuvir and velpatasvir the SVR rate was 97%, and while the adverse event rate was 50% there were only 3 severe adverse events, none of which were attributed to therapy and there were no liver related adverse events).
Pariente A, Arpurt JP, Rémy AJ, Rosa-Hézode I, Causse X, Heluwaert F, Macaigne G, et al. (2019). Association nationale des gastroentérologues des hôpitaux (ANGH). Hepatitis C treatment with all-oral direct-acting antivirals: Effectiveness and tolerance in a multicenter, prospective, observational study from French general hospitals (APROVVIE, ANGH). Presse Med. (Among 1123 patients with chronic hepatitis C treated at 24 French general hospitals with various interferon-free antiviral regimens for 12 or 24 weeks, the overall response rate was 91% with lower responses among 553 patients with cirrhosis, two of whom developed hepatic decompensation and died).
Shiha G, Esmat G, Hassany M, Soliman R, Elbasiony M, Fouad R, Elsharkawy A, et al. (2019). Ledipasvir/sofosbuvir with or without ribavirin for 8 or 12 weeks for the treatment of HCV genotype 4 infection: results from a randomised phase III study in Egypt. Gut. (Among 255 adults with chronic hepatitis C, genotype 4, [23% with cirrhosis] who were treated with ledipasvir and sofosbuvir with or without ribavirin for 12 or 24 weeks, the SVR rate ranged from 90% to 100% and adverse events in 37% to 63%, but there were no treatment related serious adverse events or reported episodes of decompensation).
Laurain A, Metivier S, Haour G, Larrey D, Dorival C, Hezode C, Zoulim F, et al., ANRS/AFEF HEPATHER study group. (2019). Safety and efficacy of the combination simeprevir-sofosbuvir in HCV genotype 1-and 4-mono-infected patients from the French ANRS CO22 hepather cohort. BMC Infect Dis. (Among 599 patients with chronic hepatitis C, genotype 1 or 4, treated between 2013 and 1018 with sofosbuvir and ledipasvir with or without ribavirin for 12 or 24 weeks in multiple French centers , the overall SVR rate was 93%, which was somewhat lower in patients with cirrhosis [91%] among whom adverse events were more frequent but there was no mention of decompensation during therapy).
Mangia A, Piazzolla V, Giannelli A, Visaggi E, Minerva N, Palmieri V, Carraturo I, et al. (2019). SVR12 rates higher than 99% after sofosbuvir/velpatasvir combination in HCV infected patients with F0-F1 fibrosis stage: A real world experience. PLoS One. (Among 1319 patients with chronic hepatitis C, genotypes 1,2,3,4 and 6, treated with sofosbuvir and ledipasvir for 12 weeks enrolled in a Italian registry, the SVR rate was 98.5% and was 98% in 282 with cirrhosis and four patients died with decompensated cirrhosis).
Naggie S, Fierer DS, Hughes MD, Kim AY, Luetkemeyer A, Vu V, Roa J, et al. (2019). Acquired Immunodeficiency Syndrome Clinical Trials Group (ACTG) A5327 Study Team. Ledipasvir/sofosbuvir for 8 weeks to treat acute hepatitis C virus infections in men with human immunodeficiency virus infections: Sofosbuvir-containing regimens without interferon for treatment of acute HCV in HIV-1 infected individuals. Clin Infect Dis. (Among 27 HIV positive men with acute hepatitis C treated with sofosbuvir and ledipasvir for 8 weeks, all achieved an SVR and there were no treatment related serious adverse events).
Borgia SM, Dearden J, Yoshida EM, Shafran SD, Brown A, Ben-Ari Z, Cramp ME, et al. (2019). Sofosbuvir/velpatasvir for 12 weeks in hepatitis C virus-infected patients with end-stage renal disease undergoing dialysis. J Hepatol. (Among 59 patients with chronic hepatitis C and end-stage renal disease on hemo- or peritoneal-dialysis treated with sofosbuvir and velpatasvir for 12 weeks, the SVR rate was 95% and there were no treatment related serious adverse events or hepatic adverse events).
Wahid B. (2019). Hepatotoxicity and virological breakthrough of HCV following treatment with sofosbuvir, daclatasvir, and ribavirin in patients previously treated for tuberculosis. J Med Virol. (A 71 year old man with chronic hepatitis C and decompensated cirrhosis being treated with sofosbuvir, daclatasvir and ribavirin developed virologic breakthrough and worsening ascites after 3 months of therapy).
Degasperi E, Spinetti A, Lombardi A, Landonio S, Rossi MC, Pasulo L, Pozzoni P, et al., NAVIGATORE-Lombardia and Veneto Study Groups. (2019). Real-life effectiveness and safety of sofosbuvir/velpatasvir/ voxilaprevir in hepatitis C patients with previous DAA failure. J Hepatol. (Among 179 patients with chronic hepatitis C receiving the combination of sofosbuvir, velpatasvir and voxilaprevir for 12 weeks after failure of previous direct acting agents in 27 Northern Italian centers, the SVR rate was 91% overall, 25% developed adverse events, which were serious in 6%, but none were considered treatment related and none were liver related).
Rosenthal P, Schwarz KB, Gonzalez-Peralta RP, Lin CH, Kelly DA, Nightingale S, Balistreri WF, et al. (2020). Sofosbuvir and ribavirin therapy for children aged 3 to <12 years with hepatitis C virus genotype 2 or 3 infection. Hepatology. (Among 54 children, ages 3 to 12 years, with chronic hepatitis C genotypes 2 and 3 treated with sofosbuvir and ribavirin for 12 or 24 weeks, the SVR rate was 98% and there were no serious adverse events related to sofosbuvir).
Schwarz KB, Rosenthal P, Murray KF, Honegger JR, Hardikar W, Hague R, Mittal N, et al. (2020). Ledipasvir-sofosbuvir for 12 weeks in children 3 to <6 years old with chronic hepatitis C. Hepatology. (Among 34 children, ages 3 to 6 years, with chronic hepatitis C, genotypes 1 and 4, the SVR rate was 97% and there were no serious adverse events or laboratory abnormalities).
Gheorghe LS, Preda C, Iliescu L, Istratescu D, Chifulescu AE, Pop CS, Trifan A, et al. (2020). Efficacy and safety of ledispavir/sofosbuvir with or without ribavirin in patients with decompensated liver cirrhosis and hepatitis C infection: a cohort study. J Gastrointestin Liver Dis. (Among 349 patients with chronic hepatitis C and decompensated cirrhosis who were treated with sofosbuvir and ledipasvir with or without ribavirin for 12 or 24 weeks, the overall SVR rate was 85% and serious adverse events occurred in 5% which were severe decompensation events in 2.6%).
Atsukawa M, Tsubota A, Kondo C, Toyoda H, Nakamuta M, Takaguchi K, Watanabe T, et al., KTK49 Liver Study Group. (2020). Real-world clinical application of 12-week sofosbuvir/velpatasvir treatment for decompensated cirrhotic patients with genotype 1 and 2: a prospective, multicenter study. Infect Dis Ther. (Among 71 Japanese patients with chronic hepatitis C and cirrhosis [Child Class A in 4, B in 47, and C in 17] treated with sofosbuvir and velpatasvir for 12 weeks, the SVR rate was 94% and two patients had to discontinue therapy early because of severe adverse events, cholecystitis and one variceal hemorrhage).
Takaoka Y, Miura K, Morimoto N, Ikegami T, Kakizaki S, Sato K, Ueno T, et al., Liver Investigators in the Northern Kanto Study (LINKS) group. (2021). Real-world efficacy and safety of 12-week sofosbuvir/velpatasvir treatment for patients with decompensated liver cirrhosis caused by hepatitis C virus infection. Hepatol Res. (Among 72 patients with chronic hepatitis C and decompensated cirrhosis [Class B 59, Class C 13] treated with sofosbuvir and velpatasvir for 12 weeks, the SVR rate was 96%, but only 75% improved clinically, worsening of Child class to C [2%], and adverse events including hepatic encephalopathy in 11 [15%]).
Baatarkhuu O, Lee JS, Amarsanaa J, Kim DY, Ahn SH, Naranzul N, Enkhtuya D, et al. (2021). Efficacy and safety of ledipasvir/sofosbuvir in 5,028 Mongolian patients infected with genotype 1 hepatitis C virus: A multicenter study. Clin Mol Hepatol. (Among 5025 Mongolian patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir for 12 weeks between 2016 and 2020 as a part of a nationwide program for elimination of hepatitis C, the SVR rate was 99% and there were no severe adverse events).
Peters MG, Kottilil S, Terrault N, Amara D, Husson J, Huprikar S, Florman S, et al. (2021). Retrospective-prospective study of safety and efficacy of sofosbuvir-based direct-acting antivirals in HIV/HCV-coinfected participants with decompensated liver disease pre- or post-liver transplant. Am J Transplant. (Among 68 patients with chronic hepatitis and C and HIV infection with cirrhosis and end-stage liver disease treated with sofosbuvir-based all oral therapy, the SVR rate in those treated post-liver transplant was 95% [25/26] and 90% [38/42] pre-transplant and while severe adverse events were frequent, no patient had to discontinue therapy early because of side effects).
Terrault NA, Burton J, Ghobrial M, Verna E, Bayer J, Klein C, Victor D, et al. (2021). Prospective multicenter study of early antiviral therapy in liver and kidney transplant recipients of HCV-viremic donors. Hepatology. (Among 24 patients receiving an HCV RNA positive liver [n=13] or renal [n=11] transplant who were treated shortly after documentation of infection with sofosbuvir and velpatasvir for 12 weeks, all with follow up achieved an SVR).
Matthews GV, Bhagani S, Van der Valk M, Rockstroh J, Feld JJ, Rauch A, Thurnheer C, et al., REACT study group. (2021). Protocol Steering Committee; Coordinating Centre; Site Principal Investigators. Sofosbuvir/velpatasvir for 12 vs. 6 weeks for the treatment of recently acquired hepatitis C infection. J Hepatol. (Among 188 patients with recently acquired HCV infection treated with sofosbuvir and velpatasvir for 6 or 12 weeks, SVR rates were 82% vs 91%, and adverse events were generally mild, none resulting in early discontinuation and with only one serious adverse event thought to be treatment related: self-limited rhabdomyolysis that resolved despite continuing therapy).
Tada T, Kurosaki M, Nakamura S, Hasebe C, Kojima Y, Furuta K, Kobashi H, et al. (2021). Real-world clinical outcomes of sofosbuvir and velpatasvir treatment in HCV genotype 1- and 2-infected patients with decompensated cirrhosis: A nationwide multicenter study by the Japanese Red Cross Liver Study Group. J Med Virol. (Among 65 Japanese adults with chronic hepatitis C and decompensated cirrhosis treated with sofosbuvir and velpatasvir for 12 weeks, the SVR rate was 92% and there were no serious adverse event rates).
El Kassas M, Abdeen N, Omran D, Alboraie M, Salaheldin M, Eltabbakh M, Farghaly R, et al. (2021). Safety and efficacy of sofosbuvir/ledipasvir and sofosbuvir/daclatasvir in the treatment of hepatitis C in patients with decompensated cirrhosis. Eur J Gastroenterol Hepatol. (Among 145 Egyptian patients with chronic hepatitis C and decompensated cirrhosis treated with sofosbuvir combined with ledipasvir or daclatasvir, the SVR rate was 88% and 11 patients had to discontinue therapy early because of ALT elevations or worsening decompensation).
Cheng PN, Mo LR, Chen CT, Chen CY, Huang CF, Kuo HT, Lo CC, et al., TACR investigators. (2022). Sofosbuvir/velpatasvir for hepatitis C virus infection: real-world effectiveness and safety from a nationwide Registry in Taiwan. Infect Dis Ther. (Among 3480 patients with chronic hepatitis C [15% with cirrhosis] treated with sofosbuvir and velpatasvir with or without ribavirin in a Taiwan national registry, the SVR rate was 99%, and adverse event rate 10%. only 0.6% rated as serious, while 0.3% had ALT elevations above 5 times ULN).

## OTHER REFERENCE LINKS

1 Recent References on Sofosbuvir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Sofosbuvir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Sofosbuvir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sofosbuvir)